# Azathioprine

## OVERVIEW

### Introduction

Azathioprine is a purine analogue and prodrug of mercaptopurine that is used as an immunosuppressive agent in organ transplantation to prevent rejection and in autoimmune diseases as a corticosteroid sparing agent. Azathioprine is associated with minor, usually transient and asymptomatic elevations in serum aminotransferase levels during therapy and with rare instances of acute, cholestatic liver injury and, with long term use, noncirrhotic portal hypertension as a result of nodular regenerative hyperplasia or sinusoidal obstruction syndrome.

### Background

Azathioprine (ay" za thye' oh preen) is an imidazolyl derivative and prodrug of mercaptopurine that inhibits lymphocyte function by antagonism of purine metabolism, thus inhibiting DNA, RNA and subsequent protein synthesis. Azathioprine inhibits the maturation of T cells and blocks delayed hypersensitivity reactions; it also has antiinflammatory activity. Azathioprine was introduced into use in the early 1960s and represented a major breakthrough in the development of antirejection therapy, allowing for more widespread and successful use of kidney, heart and liver transplantation. Azathioprine was approved for use in the United States in 1968 and is still widely used in transplantation and in treatment of autoimmune conditions such as Crohn disease, rheumatoid arthritis and autoimmune hepatitis. Azathioprine is available generically and under the brand name of Imuran as tablets of 50, 75 and 100 mg; a parenteral formulation is also available. The usual dose is 1 to 3 mg per kilogram or 50 to 150 mg daily and it is typically given long term. Common side effects include nausea, abdominal upset, rash, aphthous ulcers and dose related bone marrow suppression. Long term use of azathioprine is associated with an increased risk for malignancy, including lymphoma and possibly hepatocellular carcinoma.

### Hepatotoxicity

Azathioprine has been associated with several forms of hepatotoxicity, including mild, transient and asymptomatic rises in serum aminotransferase levels, an acute cholestatic injury developing during the first year of starting therapy, and a chronic hepatic injury marked by peliosis hepatis, veno-occlusive disease or nodular regenerative hyperplasia that typically arises 1 to 5 years after starting azathioprine.

Mild serum aminotransferase elevations can occur during azathioprine therapy, particularly with high doses during the first 12 weeks of therapy. These elevations are generally asymptomatic, benign and self-limited, resolving rapidly either with stopping therapy and often even with continuing treatment at a lower dose. ALT elevations during azathioprine therapy may be due to a direct toxic effect of the drug; ALT elevations as well as myelotoxicity have been linked to higher levels of methyl-mercaptopurine, a product of one of the metabolic pathways of azathioprine metabolism.

Azathioprine can also cause an acute, clinically apparent liver injury that is typically cholestatic. This complication is uncommon but not rare, occurring in less than one in a thousand treated patients, with estimates ranging from 1:333 to 1:1,300 exposed persons. The acute cholestatic injury due to azathioprine usually presents with fatigue and jaundice after 2 to 12 months of starting therapy. The serum ALT and alkaline phosphatase tend to be only mildly or moderately elevated and in a mixed cholestatic-hepatocellular pattern. Rash, fever and eosinophilia are uncommon and autoantibodies are generally not found. Liver biopsy typically shows intrahepatic cholestasis with focal hepatocellular necrosis and scant inflammation suggestive of a cholestatic hepatitis. In some cases, the injury resembles the "bland cholestasis" as occurs with estrogens or anabolic steroids. Indeed, azathioprine induced cholestasis resembles idiopathic cholestasis of pregnant and may precipitate or exacerbation that condition in women who are The liver injury usually resolves rapidly on stopping, but prolonged cholestasis has been reported and some cases have been associated with vanishing bile duct syndrome, which can be progressive and eventually fatal. This form of azathioprine hepatotoxicity appears to be idiosyncratic and, with other nonhepatic hypersensitivity reactions (fever, rash, vasculitis), is possibly linked to the nitroimidazole component of azathioprine.

Azathioprine, like other thiopurines, can also cause chronic liver injury and long term therapy has been linked to the development of portal hypertension and nodular regenerative hyperplasia. This form of chronic azathioprine hepatotoxicity typically presents with fatigue and signs and symptoms of portal hypertension accompanied by mild liver enzyme abnormalities and minimal jaundice arising 6 months to many years after starting azathioprine. Liver biopsy shows nodular regenerative hyperplasia and varying amounts of sinusoidal dilation and central vein injury. This syndrome can progress to hepatic failure, particularly if azathioprine is continued, but clinical improvement after stopping therapy is typical. The onset of this syndrome may be acute with abdominal pain and ascites, in which situation liver biopsy usually shows sinusoidal dilation, central congestion and injury to sinusoidal endothelial cells suggestive of veno-occlusive disease which is currently referred to as sinusoidal obstructive syndrome. Typically, serum aminotransferase levels and alkaline phosphatase levels are minimally elevated, even in the presence of hyperbilirubinemia and other manifestations of hepatic dysfunction and portal hypertension (thrombocytopenia).

Finally, long term therapy with azathioprine and other thiopurines has been implicated in leading to the development of malignancies, including hepatocellular carcinoma (HCC) and hepatosplenic T cell lymphoma (HSTCL). Both of these complications are rare, but have been reported in several dozen case reports and small case series. In neither instance has the role of thiopurine therapy in causing the malignancies been proven, and similar cases have been described in patients with autoimmune conditions or after solid organ transplantation who have not received thiopurines. Hepatocellular carcinoma typically arises after years of azathioprine or mercaptopurine therapy and in the absence of accompanying liver disease (although sometimes with focal hepatic glycogenosis). The HCC is most frequently found on an imaging study done of an unrelated condition. The prognosis is more favorable than that of HCC associated with cirrhosis. Hepatosplenic T cell lymphoma has been reported largely among young men with inflammatory bowel disease and long term immunosuppression with a thiopurine, with or without anti-tumor necrosis factor therapy. The typical presentation is with fatigue, fever, hepatosplenomegaly and pancytopenia. The diagnosis is made by bone marrow or liver biopsy showing marked infiltration with malignant T cells. HSTCL is poorly responsive to antineoplastic therapy and has a high mortality rate.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Histopathology

The typical histologic pattern of acute liver injury caused by azathioprine is a cholestatic hepatitis with mild parenchymal injury and inflammation, presence of bile plugs in canaliculi and portal inflammation with chronic inflammatory cells. In some instances there is bile duct injury and cholestasis can be prolonged.

CHOLESTATIC HEPATITIS (EXAMPLE 1)

| This case shows cholestatic hepatitis due to azathioprine. In zone 3 there was hepatocellular and canalicular (arrows) cholestasis. Foamy macrophages containing bile pigment fill the sinuses. The dark red line through the photo is an artifactual fold in the tissue on the glass microscope slide.
| The portal areas showed a mild, predominantly lymphocytic infiltrate associated with mild bile duct injury. The positions of ducts (D) and arteries (A) are indicated.

### CHOLESTATIC HEPATITIS (EXAMPLE 2)

| This case also shows a very mild cholestatic hepatitis, similar to example 1. A large bile plug (arrow) can be seen near the central vein (V) in this photo.
| A mild lymphocytic infiltrate was seen in some of the portal areas. Hepatocytes in this case have pale staining cytoplasm consistent with glycogenosis. The location of bile ducts (D) is indicated for orientation.

### Mechanism of Injury

Azathioprine is a pro-drug of mercaptopurine and the mechanism of liver injury is probably similar to that of mercaptopurine. Both drugs appear to have some degree of direct hepatotoxicity which has been demonstrated in dogs that are very sensitive to its toxicity. Azathioprine undergoes extensive hepatic metabolism, first to 6-mercaptopurine and thereafter to other thiopurines via at least 3 different pathways. Patients with high levels in thiopurine methyltransferase may have a higher rate of hepatotoxicity while low levels may predispose to bone marrow suppression. Thus, hepatotoxicity is often accompanied by low or modest levels of the active metabolite, 6-thioguanine nucleotide (6-TGN) and high levels of the toxic metabolite, methylmercaptopurine nucleotide (MMPN). The cholestatic liver injury from azathioprine and mercaptopurine, however, appears to have a different pathogenesis and may be dose independent and immunologically mediated. The similarity of azathioprine cholestatic injury to idiopathic cholestasis of pregnancy suggests that inhibition of biliary transporters may be involved. The cause of the nodular regenerative hyperplasia that develops after long term azathioprine therapy is not well defined, but it appears to be due to injury to endothelial cells that causes variable degrees of venous outflow obstruction or portal venopathy and vascular damage that promote the nodular transformation.

### Outcome and Management

Both the acute cholestasis and the chronic nodular regeneration caused by azathioprine improve upon stopping the medication, but instances of progression to hepatic failure despite discontinuation of azathioprine have been reported with both syndromes. There are no known specific treatments for azathioprine hepatotoxicity. Rechallenge with azathioprine usually results in recurrence of the injury (within days to weeks) and should be avoided. Some patients have tolerated switching therapy to mercaptopurine or thioguanine, but substitution with a structurally unrelated immunosuppressive agent is more appropriate.

Drug Class: Antineoplastic Agents, Antirheumatic Agents, Transplant Drugs, Purine Analogues; Gastrointestinal Agents

book-part://Transplant_Drugs/Other Drugs in the Subclass, Purine Analogues/Thiopurines: Mercaptopurine, Thioguanine

## CASE REPORTS

### Case 1. Acute cholestatic hepatitis due to azathioprine.(1)

A 22 year old man with systemic lupus erythematosus with polyserositis and nephritis was started on high doses of prednisone to which azathioprine was added in an initial doses of 50 mg daily, later increasing to 100 mg daily. Three weeks later, serum ALT and alkaline phosphatase levels, which had been normal, began to rise and a week later he became jaundiced (Table). Physical examination showed no evidence of chronic liver disease. Tests for hepatitis A and B and CMV infection were negative. Serum autoantibodies had decreased during the month of immunosuppressive therapy. Azathioprine was stopped promptly, but liver tests worsened for the next week. A liver biopsy showed marked cholestasis and centrolobular ballooning degeneration with an occasional acidophil body, but scant inflammation and no fibrosis. Liver tests subsequently began to improve and were normal 6 weeks later.

#### Key Points

Medication: | Azathioprine (50→100 mg daily)
Pattern: | Mixed (R=4.8 initially, falling to 1.8)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3.5 weeks
Recovery: | 6 weeks
Other medications: | Prednisone, clonidine (0.2 mg twice daily); both continued

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Direct Bilirubin* (mg/dL) | Other
0 | | 25 | 75 | 0.0
1 week | | 105 | 80 | 0.2
3 weeks | | 110 | 90 | 0.1
3.2 weeks | 0 | 705 | 290 | 1.2 | Admission
4.5 weeks | 1 week | 530 | 550 | 4.8 | Liver biopsy
6 weeks | 3 weeks | 350 | 410 | 0.2
7 weeks | 4 weeks | 180 | 290 | 0.3
9 weeks | 6 weeks | 40 | 95 | 0.1
Normal Values | | <50 | <100 | <0.3

* Estimated from Figure 1.

#### Comment

This is a typical case of acute idiosyncratic liver injury caused by azathioprine. The initial serum enzyme pattern was indicative of mixed hepatocellular-cholestatic injury, but subsequently values were indicative of cholestatic hepatitis, which was supported by the finding of marked cholestasis with minimal inflammation by liver biopsy. The clinical course and presentation may have been altered by the concurrent use of high doses of prednisone (perhaps accounting for lack of eosinophils on liver biopsy). This syndrome appears to be more common with higher doses of azathioprine.

### Case 2. Nodular regenerative hyperplasia during long term azathioprine therapy after renal transplantation.(2)

A 33 year old man underwent renal transplantation for end-stage kidney disease due to Goodpasture’s syndrome. After a single episode of rejection, he was maintained on prednisolone (20 mg daily) and high doses of azathioprine (3 mg/kg daily). His liver tests were normal before transplantation, but began to rise approximately 15 months afterwards (Table). Hepatitis serology was negative and autoantibodies were not detected. He maintained good renal function. Two years after transplant he was found to have an enlarged liver and spleen and ascites. A liver biopsy showed nodular regenerative hyperplasia with minimal fibrosis and scant inflammation. Ascites was controlled with diuretics.

#### Key Points

Medication: | Azathioprine (3 mg/kg/day)
Pattern: | Cholestatic (R=0.9)
Severity: | 4+ (symptoms and ascites)
Latency: | 15 months
Recovery: | Unclear
Other medications: | Prednisolone

#### Laboratory Values

Time After Transplant | AST (U/L) | Alk P (U/L) | GGT (U/L) | Bilirubin (mg/dL) | Other
6 months | 18 | 96 | 18 | 0.5
15 months | 21 | 77 | 45 | 0.4
21 months | 56 | 185 | 240 | 2.1
27 months | 58 | 143 | 183 | 2.0 | Ascites: biopsy
35 months | 42 | 136 | 168 | 2.0
Normal | <40 | <115 | <31 | <1.2

#### Comment

Nodular regenerative hyperplasia appears to be the result of vascular injury, either to endothelial cells lining the sinusoids or portal veins responsible for venous inflow. The liver responds with regenerative changes that alter the structure of the liver, producing nodules with varying sizes of hepatocytes and resultant portal hypertension. Liver tests are generally minimally abnormal and signs of portal hypertension arise (ascites, esophageal varices) that appear to indicate the presence of cirrhosis, but liver biopsy shows little or no fibrosis and superficially may appear normal. A reticulin stain of elastic fibers, however, usually demonstrates nodularity of the liver. Patients with nodular regeneration can develop hepatic decompensation, particularly in response to variceal hemorrhage, hemodynamic instability, bacterial peritonitis or septicemia. All of the thiopurines (azathioprine, thioguanine and mercaptopurine) have been associated with the development of nodular regenerative hyperplasia. This example demonstrates the silent nature of its onset and the challenge in its diagnosis. An early clue to the development of portal hypertension is a gradual decrease in platelet count, even while still in the normal range. The current case report did not make clear whether azathioprine was stopped, but other reports have indicated that patients often improve clinically with discontinuation of the implicated medication.

### Case 3. Nodular regenerative hyperplasia during azathioprine therapy for inflammatory bowel disease.(3)

A 44 year old man with severe ulcerative colitis requiring long term corticosteroid therapy was started on azathioprine (2.5 mg/kg/day) and was found to have developed mild liver test abnormalities six months later. Serum aminotransferase, alkaline phosphatase and gamma glutamyl transpeptidase (GGT) levels were 1.1 to 1.7 times the upper limit of normal (ULN). Serum bilirubin and prothrombin time were normal and all tests for viral hepatitis and autoimmune markers were negative. The platelet count had fallen from normal to 129,000/μL. Hepatic imaging using magnetic resonance and ultrasound were normal. Endoscopy did not reveal esophageal varices or portal hypertensive gastropathy. A liver biopsy, however, showed early changes of nodular regenerative hyperplasia, with scant inflammation and no evidence of injury to central veins or bile ducts. During the ensuing 6 to 9 months, serum GGT levels continued to rise, and eventually azathioprine was stopped. Subsequently, GGT levels fell gradually and the platelet count stabilized. The patient remained asymptomatic of liver disease, and subsequently the ulcerative colitis was adequately controlled with corticosteroids only.

#### Key Points

Medication: | Azathioprine (200 mg/day for 16 months)
Pattern: | Cholestatic (R=0.9)
Severity: | 1+ (asymptomatic liver test abnormalities)
Latency: | 6 months
Recovery: | Unclear
Other medications: | Prednisolone

#### Laboratory Values

Time After Transplant | Time After Stopping | GGT (times ULN) | Platelets (1000/μL) | Other
0 | | 1.0 | 320
6 months | | 1.1 | 129
1 year | 0 | 10.2 | 110
1.5 years | 6 months | 9.0 | 145
2 years | 1 year | 7.2 | 110
2.5 years | 1.5 years | 5.9 | 110
3 years | 2 years | 1.5 | 150
Normal Values | | <31 | >160

#### Comment

Nodular regenerative hyperplasia can arise fairly rapidly during long term therapy with thiopurines such as azathioprine. The condition is largely asymptomatic, but clues to its presence include mild liver test abnormalities (particularly GGT) and a fall in platelet count. Imaging usually demonstrates enlargement of the spleen and mild abnormalities in the appearance of the liver. With progression of nodular transformation, portal hypertension can arise and distinct hepatic decompensation can occur as a complication of incurrent infections, variceal hemorrhage or renal failure.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Azathioprine – Generic, Imuran®

DRUG CLASS

Antineoplastic Agents

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Azathioprine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Azathioprine | 446-86-6 | C9-H7-N7-O2-S
Mercaptopurine | 6112-76-1 | C5-H4-N4-S.H2-O
Thioguanine | 154-42-7 | C5-H5-N5-S

The thiopurines include azathioprine, mercaptopurine and thioguanine, all of which are sulphur substituted purine bases. The prototype of this class is mercaptopurine which was introduced into clinical medicine in the 1950's, largely as an antineoplastic agent. Azathioprine was developed and introduced into clinical medicine in the mid-1960's as a prodrug of mercaptopurine having a nitroimidazole attached to the sulphur of the mercaptopurine molecule. Azathioprine has been used largely as an immunosuppressive agent.

## CITED REFERENCES

1 DePinho RA, Goldberg CS, Lefkowitch JH. Azathioprine and the liver: evidence favoring idiosyncratic, mixed cholestatic-hepatocellular injury in man. Gastroenterology 1984; 86: 162-5. 6689657
2 Jones MC, Best PV, Catto GRD. Is nodular regenerative hyperplasia of the liver associated with azathioprine therapy after renal transplantation. Nephrol Dial Transplant 1988; 3: 330-3. 3140109
3 Daniel F, Cadranel JF, Seksik P, Cazier A, Duong Van Huyen JP, Ziol M, Coutarel P, et al. Azathioprine induced nodular regenerative hyperplasia in IBD patients. Gastroenterol Clin Biol 2005; 29: 600-34. 15980758

## ANNOTATED BIBLIOGRAPHY

References updated: 05 March 2026

Abbreviations used: TPMT, thiopurine methyltransferase; HSTCL, hepatosplenic T-cell lymphoma; HCC, hepatocellular carcinoma; MMPN, methylmercaptopurine nucleotides; 6-TGN, 6-thioguanine nucleotides; ICP, idiopathic cholestasis of pregnancy.

Zimmerman HJ. Antipurines. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 687-9. (Expert review of hepatotoxicity of thiopurines published in 1999).
DeLeve LD. Thiopurines. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 555-6. (Review of hepatotoxicity of thiopurines).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Purine analogues. Cytotoxic agents. In, Brunton LL, Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1184-6. (Textbook of pharmacology and therapeutics).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan D. Purine analogues. Cytotoxic agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1701-2. (Textbook of pharmacology and therapeutics).
McIlvanie SK, MacCarthy JD. Hepatitis in association with prolonged 6-mercaptopurine therapy. Blood 1959; 14: 80-90. (Four cases of acute "toxic" liver injury during mercaptopurine therapy of leukemia in children, ages 4-13 years, arising 2-6 months after starting drug [bilirubin 4.5-8.7 mg/dL, Alk P mildly elevated]). 13607581
Clark PA, Hsia YE, Huntsman RG. Toxic complications of treatment with 6-mercaptopurine: two cases with hepatic necrosis and intestinal ulceration. Br Med J 1960; 1: 393-5. (Two cases; 5 year old boy with acute leukemia developed jaundice after 7 weeks of mercaptopurine therapy [bilirubin 6.6 mg/dL, minimal Alk P elevations], on autopsy liver showed severe centrolobular hepatic necrosis; 40 year old man with acute leukemia developed jaundice after 4 weeks of mercaptopurine [bilirubin 9.5 mg/mL, ALT 140 U/L, Alk P 2 times ULN], with rapid progress and death, autopsy showing centrilobular necrosis). 13810473
Einhorn M, Davidsohn I. Hepatotoxicity of mercaptopurine. JAMA 1964; 188: 802-6. (Among 38 patients with leukemia treated with mercaptopurine, 16 developed jaundice, resolving with stopping in half and recurring in two with rechallenge; onset in 4-8 weeks [bilirubin 3.6-14.8 mg/dL, ALT 21-140 U/L, Alk P 1-6 times ULN]). 14132534
Mackay IR, Weiden S, Ungar B. Treatment of chronic active hepatitis and lupoid hepatitis with 6-mercaptopurine and azathioprine. Lancet 1964; 1: 899-902. (Experience in using mercaptopurine and azathioprine in 5 patients with autoimmune hepatitis, mentions that hyperbilirubinemia was a side effect of higher doses, resolving with dose modification). 14124080
Corley CC Jr, Lessner HE, Larsen WE. Azathioprine therapy of "autoimmune" diseases. Am J Med 1966; 41: 404-12. (Experience in using azathioprine in 46 patients with various autoimmune diseases, mostly an idiopathic thrombocytopenic purpura and lupus erythematosus; side effects including nausea and vomiting occurred with higher doses, mild cytopenias were common, and one patient had jaundice after 6 months [350 mg/day] [bilirubin 3.8 mg/L, mild Alk P and ALT elevations], biopsy showing cholestasis). 5330635
Krawitt EL, Stein JH, Kirkendall WM, Clifton JA. Mercaptopurine hepatotoxicity in a patient with chronic active hepatitis. Arch Intern Med. 1967; 120: 729-34. (18 year old girl with autoimmune hepatitis poorly controlled on prednisone developed fatigue and jaundice within 2-3 weeks of starting mercaptopurine, with worsening hepatic function, multiorgan failure and death). 4168362
Shorey J, Schenker S, Suki WN, Combes B. Hepatotoxicity of mercaptopurine. Arch Intern Med 1968; 122: 54-8. (Two cases; 45 year old man developed malaise and jaundice 4 months after starting mercaptopurine for glomerulonephritis [bilirubin 9.9 mg/dL, AST 112 U/L, Alk P 3 times ULN], resolving within 6 weeks of stopping; 39 year old woman developed jaundice 2-3 months after starting mercaptopurine [bilirubin 16.4 mg/dL, AST 314 U/L, Alk P 4 times ULN], with sudden unexplained death shortly after, autopsy showing intrahepatic cholestasis, with scant necrosis). 5659378
Lascari AD, Givier RL, Saper RT, Hill LF. Portal hypertension in a case of acute leukemia treated with antimetabolites for 10 years. N Engl J Med 1968; 279: 303-6. (6 year old girl with acute leukemia and long term chemotherapy including mercaptopurine, developed splenomegaly after 3 years with subsequent recurrent variceal hemorrhage; splenectomy and porto-caval shunt yielded excellent outcome; biopsy showing fibrosis without cirrhosis). 5301748
Robert J, Barbier P, Manaster J, Jacobs E. Hepatotoxicity of cytostatic drugs evaluated by liver function tests and appearance of jaundice. Digestion 1968; 1: 229-32. (Analysis of 417 courses of cytostatic therapy with various agents; half of patients receiving mercaptopurine developed elevations in serum bilirubin, but no specifics given). 5696244
Sparberg M, Simon N, Del Greco F. Intrahepatic cholestasis due to azathioprine. Gastroenterology 1969; 57: 439-41. (44 year old man developed jaundice 13 months after renal transplant [bilirubin 21 mg/dL, ALT 94 U/L, Alk P normal], biopsy showing cholestasis without hepatocyte necrosis; patient died after withdrawal of azathioprine and increase in corticosteroids). 4951148
Lehmann GW. [Intrahepatic cholestasis caused by 6-mercaptopurine]. Kinderarztl Prax 1969; 37: 506-11. German. PMID: 5379242 (15 year old girl with acute leukemia developed nausea followed by jaundice 2 months after starting mercaptopurine [bilirubin 10.6 rising to 38.1 mg/dL, ALT 42 U/L, Alk P ~2 times ULN, eosinophils 15%], ultimately responding to prednisolone, but subsequent relapse of leukemia).
Drinkard JP, Stanley TM, Dornfeld L, Austin RC, Barnett EV, Pearson CM, Vernier RL, et al. Azathioprine and prednisone in the treatment of adults with lupus nephritis. Medicine (Baltimore) 1970; 49: 411-32. (Report on 20 patients with lupus nephritis treated with combination of prednisone and azathioprine; hepatotoxicity occurred in one patient developing jaundice at 11 months [bilirubin 11.4 mg/dL, ALT 80 U/L and Alk P ~1.5 times ULN], resolving with stopping). 4924695
Malekzadeh MH, Grushkin CM, Wright HT Jr, Fine RN. Hepatic dysfunction after renal transplantation in children. J Pediatr 1972; 81: 279-85. (Nine of 63 children with renal transplants had evidence of liver disease, 8 considered due to azathioprine, arising 3-30 months after transplant [bilirubin 1.2-24 mg/dL, ALT 116-500 U/L, Alk P 1-10 times elevated], improving on stopping). 4339534
Zarday A, Veith FJ, Gliedman ML, Soberman R. Irreversible liver damage after azathioprine. JAMA 1972; 222: 690-1. (27 year old woman developed chronic liver disease after renal transplantation, improving on stopping azathioprine, but then progressing to end stage liver disease; in retrospect, possibly due to hepatitis C). 4562099
Millard PR, Herbertson BM, Evans DB, Calne RY. Azathioprine hepatotoxicity in renal transplantation. Transplantation 1973; 16: 527-30. Not in PubMed (Complex analysis of patients after renal transplantation finding no correlation between changes in azathioprine dose and changes in ALT levels).
Briggs WA, Lazarus JM, Birtch AG, Hampers CL, Hager EB, Merrill JP. Hepatitis affecting hemodialysis and transplant patients. Arch Intern Med 1973; 132: 21-8. (Analysis of 14 patients who developed hepatitis B while on renal dialysis and 14 after renal transplant; reinstitution of azathioprine was often associated with exacerbation of the hepatitis). 4577389
Ireland P, Rashid A, von Lichtenberg F, Cavallo T, Merrill JP. Liver disease in kidney transplant patients receiving azathioprine. Arch Intern Med 1973; 132: 29-37. (Analysis of course of liver disease in 24 kidney transplant patients suggested that azathioprine had little or no effect on course of what was likely chronic viral hepatitis in transplant patients). 4577390
Koretz RL. Azathioprine in liver disease. Arch Intern Med 1974; 133: 870-1. Replies by authors. PMID: 4595401 (Letter in response to Briggs [1973] and Ireland [1973] pointing out that the patients were from the same institution and may have been the same in the two studies, but that conclusions regarding safety of azathioprine were different).
Du Vivier A, Munro DD, Verbov J. Treatment of psoriasis with azathioprine. Br Med J 1974; 1: 49-51. (Among 29 patients with psoriasis treated with azathioprine, 2 developed cholestasis and 8 portal fibrosis as shown by liver biopsies performed before, at 6 months and then annually). 4812392
Berne TV, Chatterjee SN, Craig JR, Payne JE. Hepatic dysfunction in recipients of renal allografts. Surg Gynecol Obstet 1975; 141: 171-5. (Among 142 patients undergoing renal transplantation, 18 developed liver disease, all while on azathioprine; in 10 patients there was improvement with stopping). 168654
Ware AJ, Luby JP, Eigenbrodt EH, Long DL, Hull AR. Spectrum of liver disease in renal transplant recipients. Gastroenterology 1975; 68: 755-64. (Liver disease developed in 31 of 82 [38%] patients undergoing renal transplantation, 8 with acute self-limited disease, 2 with acute liver failure [1 due to HBV] and 21 with chronic liver injury; all received azathioprine, but no consistent effect of stopping or modifying dose in chronic cases, possibly being due to chronic hepatitis C which could not be serologically identified in 1975). 164401
Marubbio AT, Danielson B. Hepatic veno-occlusive disease in a renal transplant patient receiving azathioprine. Gastroenterology 1975; 69: 739-43. (54 year old man developed jaundice 14 months after renal transplant [bilirubin 5.1 mg/dL, AST 125 U/L, Alk P 1.5 times ULN], progressing to liver failure and death despite stopping azathioprine promptly; biopsies and autopsy showing veno-occlusive disease; patient also had hepatitis B). 1098955
Griner PF, Elbadawi A, Packman CH. Veno-occlusive disease of the liver after chemotherapy of acute leukemia. Report of two cases. Ann Intern Med 1976; 85: 578-82. (Two men with leukemia, ages 17 and 72 years, developed abdominal pain, ascites and progressive liver failure 3-4 months after starting cyclic cytotoxic therapy with multiple agents including thioguanine [initial bilirubin 1.3 and 2.5 mg/dL, AST 348 and 48 U/L, Alk P 92 and 276 U/L]; autopsies showed acute sinusoidal obstruction syndrome [veno-occlusive disease]). 1068643
Minow RA, Stern MH, Casey JH, Rodriguez V, Luna MA. Clinico-pathologic correlation of liver damage in patients treated with 6-mercaptopurine and adriamycin. Cancer 1976; 38: 1524-8. (Combination of adriamycin [50 mg/m2/day] and mercaptopurine [500 mg/m2/day] with vincristine and prednisone for acute leukemia was associated with high rate of hepatotoxicity; in 11 cases, bilirubin rising with each course with mild elevations in ALT and Alk P; liver tissue showing central cholestasis with mild hepatocellular necrosis and fatty change). 1068739
Degott C, Rueff B, Kreis H, DuBoust A, Potet F, Benhamou JP. Peliosis hepatis in recipients of renal transplants. Gut 1978; 19: 748-53. (Among 500 patients undergoing renal transplantation between 1965-75, 55 had liver biopsy, 12 of which showed peliosis hepatis [6 major; 6 minor changes], often in association with chronic hepatitis B; in major forms there was hepatomegaly and portal hypertension; hypothesized possible role of azathioprine). 355072
Nataf C, Feldmann G, Lebrec D, Degott C, Descamps JM, Rueff B, Benhamou JP. Idiopathic portal hypertension (perisinusoidal fibrosis) after renal transplantation. Gut 1979; 20: 531-7. (Two cases of young men developing esophageal varices 1.5 and 7 years after renal transplantation and azathioprine therapy with normal liver tests and liver biopsy, but perisinusoidal fibrosis found on electron microscopy, seemingly improving once azathioprine was stopped). 381128
Topley JM, Benson J, Squier MV, Chessells JM. Hepatotoxicity in the treatment of acute lymphoblastic leukaemia. Med Pediatr Oncol 1979; 7: 393-9. (Among 21 children receiving mercaptopurine for acute leukemia, most had transient ALT elevations, but liver biopsies were often normal or showed minimal changes). 296787
Ware AJ, Luby JP, Hollinger B, Eigenbrodt EH, Cuthbert JA, Atkins CR, Shorey J, et al. Etiology of liver disease in renal-transplant patients. Ann Intern Med 1979; 91: 364-71. (Analysis of 72 episodes of liver disease occurring in 62 of 120 renal transplant recipients; 4 episodes of acute cholestasis were attributed to azathioprine, resolving with stopping or dose reduction; azathioprine did not seem to account for cases of chronic liver injury, responses to stopping being equivocal). 224742
Stromeyer FU, Ishak KG. Nodular transformation (nodular regenerative hyperplasia) of the liver. A clinicopathological study of 30 cases. Hum Pathol 1981; 1: 60-71. (30 cases of nodular regenerative hyperplasia from the files of the Armed Forces Institute of Pathology; ages 14-80 years, half males, 18 discovered incidentally, 84% splenomegaly, 58% ascites, half died, 3 with liver failure, mild elevations in AST and Alk P levels were typical; 6 had rheumatologic disorder, 7 hematologic disease; 10 on corticosteroids, several on azathioprine; detailed description of histological changes). 7203455
Whisnant JK, Pelkey J. Rheumatoid arthritis: treatment with azathioprine (IMURAN(R)). Clinical side-effects and laboratory abnormalities. Ann Rheum Dis 1982; 41 Suppl 1: 44-7. (Review of literature on 542 patients in 24 studies given azathioprine for up to 4 years; leucopenia in 26%, gastrointestinal complaints in 19%; only two reports of hepatotoxicity). 7065742
Weitz H, Gokel SM, Loeschke K, Possinger K, Eder M. Venoocclusive disease of the liver in patients receiving immunosuppressive therapy. Virchows Arch [1] 1982; 395: 245-56. PMID: 7051531 (Four cases of sinusoidal obstruction syndrome in 34-41 year old men who developed mild jaundice 9-21 months after renal transplantation [bilirubin 2.8-3.7 mg/dL, ALT 17-60 U/L, Alk P 108-673 U/L], ultimately with fatal outcomes).
D'Cruz CA, Wimmer RS, Harcke HT, Huff DS, Naiman JL. Veno-occlusive disease of the liver in children following chemotherapy for acute myelocytic leukemia. Cancer 1983; 52: 1803-7. (Three children [2 girls and 1 boy, ages 4, 8 and 14] developed sinusoidal obstruction syndrome 5-6 months after starting chemotherapy for leukemia, presenting with abdominal pain and hepatomegaly [bilirubin 1.2-2.0 mg/dL, ALT and Alk P normal], improving on decreasing dose of chemotherapy). 6578867
Harvey C, Dixon JS, Bird HA. Serum IgA concentration and hepatotoxicity in rheumatoid arthritis treated with azathioprine. Br Med J (Clin Res Ed) 1983; 287: 534. (Among 27 patients with rheumatoid arthritis treated with azathioprine [1.5 mg/kg/day], 4 developed ALT elevations 2-8 weeks after starting, all 4 had low levels of IgA before starting [mean=109 mg/dL]). 6411213
DePinho RA, Goldberg CS, Lefkowitch JH. Azathioprine and the liver: evidence favoring idiosyncratic, mixed cholestatic-hepatocellular injury in man. Gastroenterology 1984; 86: 162-5. (22 year old man with lupus erythematosus developed jaundice 3 weeks after starting azathioprine [peak direct bilirubin ~4.9 mg/dL, ALT ~710 U/L, Alk P ~560 U/L], resolving within 6 weeks of stopping; biopsy showed intrahepatic cholestasis with scant inflammation and necrosis: Azathioprine Case 1). 6689657
Eisenhauer T, Hartmann H, Rumpf KW, Helmchen U, Scheler F, Creutzfeldt W. Favorable outcome of hepatic veno-occlusive disease in a renal transplant patient receiving azathioprine, treated by portacaval shunt: report of a case and review of the literature. Digestion 1984; 30: 185-90. (45 year old man developed ascites and abdominal pain 2 years after renal transplant while on azathioprine, biopsy showing veno-occlusive disease and ascites responding to stopping azathioprine and portacaval shunt). 6389237
Watanabe A, Obata T, Nagashima H, Sakagami K, Orita K. Nonicteric liver damage with a gamma-glutamyl transpeptidase level of 5,609 units/l in a renal-transplant recipient receiving azathioprine. Acta Med Okayama 1984; 38: 533-9.6151783
Gerlag PG, Labatty S, Driessen WM, Deckers PFL, Van Hooff JP, Schroder E, Assmann KM, et al. Hepatic sinusoidal dilatation with portal hypertension during azathioprine treatment after kidney transplantation. J Hepatol 1986; 1: 339-48. (3 patients developed evidence of portal hypertension 16-24 months after renal transplant on azathioprine therapy without portal fibrosis, improvement on stopping but residual changes found during follow up). 3902952
Read AE, Wiesner RH, La Brecque DR, Tifft JG, Mullen KD, Sheer RL, Petrelle M, et al. Hepatic veno-occlusive disease associated with renal transplantation and azathioprine therapy. Ann Intern Med 1986; 104: 651-6. (Four patients with veno-occlusive disease and signs of portal hypertension 0.5-9 years after renal transplantation while on azathioprine; one improved, 3 had progressive problems with portal hypertension and hepatic failure). 3008617
Lemarchand P, Desrumeaux B, Bercoff E, Manchon ND, Chassagne P, Deshayes P, Hémet J, Bourreille J. [Cholestasis and sinusoidal dilatation following treatment with azathioprine]. Gastroenterol Clin Biol 1986; 10: 853-4. French. PMID: 3803830 (53 year old woman with rheumatoid arthritis developed jaundice 6 months after starting azathioprine [bilirubin 12.9 mg/dL, ALT 75 U/L, Alk P 1150 U/L], resolving within 1 month of stopping and relapsing 3 days after rechallenge, biopsy showed sinusoidal dilatation and intrahepatic cholestasis with minimal inflammation).
Kissel JT, Levy RJ, Mendell JR, Griggs RC. Azathioprine toxicity in neuromuscular disease. Neurology 1986; 36: 35-9. (Retrospective review of 64 patients with autoimmune neuromuscular disease treated with azathioprine for 0.5 to 16 years; dose modification for toxicity was done in 42%, most commonly for leucopenia, hepatotoxicity occurred in 9%, arising within 1-8 weeks, resolving within 1-2 months in all; recurrence on rechallenge within days). 3941781
Katzka DA, Saul SH, Jorkasky D, Sigal H, Reynolds JC, Soloway RD. Azathioprine and hepatic venoocclusive disease in renal transplant patients. Gastroenterology 1986; 90: 446-54. (3 men, ages 37-59 years, developed liver test abnormalities [bilirubin 1.5-3.5 mg/dL, ALT 44-86 U/L, Alk P 505-648 U/L] 12-32 months after starting azathioprine, 2 dying and one surviving with improvement after stopping azathioprine; all had nodular regenerative hyperplasia and sinusoidal obstructive changes on biopsy or autopsy). 3510146
Cooper C, Cotton DW, Minihane N, Cawley MI. Azathioprine hypersensitivity manifesting as acute focal hepatocellular necrosis. J R Soc Med 1986; 79: 171-3. (58 year old man with rheumatoid arthritis developed jaundice 2 weeks after starting azathioprine [bilirubin 2.3 mg/dL, ALT >300 U/L, Alk P 898 U/L], liver biopsy showing nonspecific changes and symptoms, resolving within 1 week and laboratory abnormalities within 1 month of stopping). 3701755
Barrowman JA, Kutty PK, Mu RA, Huang SN. Sclerosing hepatitis and azathioprine. Dig Dis Sci 1986; 31: 221-2. (35 year old man treated with azathioprine for 8 years developed jaundice [bilirubin 10 mg/dL, AST 350 U/L, Alk P 287 U/L], which progressed to end-stage liver disease and death 5 months later despite stopping azathioprine; clinical course possibly representing vanishing bile duct syndrome). 3943451
Adler M, Delhaye M, Deprez C, Hardy N, Gelin M, DePauw L, Vererstraeten P, et al. Hepatic vascular disease after kidney transplantation: report of two cases and review of the literature. Nephrol Dialysis Transplant 1987; 2: 183-8. (Two men, ages 31 and 40 years, developed portal hypertension due to azathioprine 9 and 4 years after kidney transplant, presenting with fatigue and abdominal distension with mild jaundice and minimal elevations in Alk P and ALT, biopsy showed changes of peliosis and sinusoidal obstruction syndrome; subsequently both had hepatic decompensation and one died). 3114679
Tage-Jensen U, Schlichting P, Thomsen HF, Høybye G, Thomsen AC. Malignancies following long-term azathioprine treatment in chronic liver disease. A report from the Copenhagen Study Group for Liver Diseases. Liver 1987; 7: 81-3. (Among 154 patients with chronic hepatitis treated with prednisone or azathioprine for an average of 7 years, all cause mortality was similar, but there were more deaths from malignancies in the azathioprine [n=13] than the prednisone [n=4] treated group; no denominator of number of patients or patient-years provided). 3613879
Gruber S, Dehner LP, Simmons RL. De novo hepatocellular carcinoma without chronic liver disease but with 17 years of azathioprine immunosuppression. Transplantation 1987; 43: 597-600. (38 year old man, with 7 year history of renal transplantation and azathioprine therapy, developed unresectable HCC despite having a noncirrhotic liver). 3033852
Fonseca V, Havard CW. Portal hypertension secondary to azathioprine in myasthenia gravis. Postgrad med J 1988; 64: 950-2. (52 year old man with myasthenia was found to have splenomegaly 3 years after starting azathioprine [150 mg/day] [bilirubin 4.1 mg/dL, AST 40 U/L, Alk P 107 U/L, platelets 103,000/ μL], biopsy showing nodular regenerative hyperplasia, with improvement in liver tests [bilirubin 1.2 mg/dL] upon stopping). 3256814
Haboubi MB, Hiam H, Whitwell HL, Ackrill P. Role of endothelial cell injury in the spectrum of azathioprine-induced liver disease after renal transplant: light microscopy and ultrastructural observations. Am J Gastroenterol 1988; 83: 256-61. (3 cases, men, ages 26-44 developing hepatomegaly and signs of portal hypertension 1-5 years after renal transplant on azathioprine; biopsies showed peliosis and nodular regenerative hyperplasia, 1 died of hepatic failure, 2 improved on stopping azathioprine; suggested endothelial cell injury). 3278593
Buffet C, Cantarovitch M, Pelletier G, Fabre M, Martin E, Charpentier B, Etienne JP, et al. Three cases of nodular regenerative hyperplasia of the liver following renal transplantation. Nephrol Dial Transplant 1988; 3: 327-30. (Three men, ages 22, 29 and 50 years, developed nodular regenerative hyperplasia with hepato-splenomegaly 24-30 months after renal transplant while on azathioprine, two had peliosis and one sinusoidal obstruction syndrome; minimal liver test abnormalities in two; jaundice in the third who had a fatal outcome [initial bilirubin 5.8 mg/dL, AST 35 U/L, Alk P 80 U/L]). 3140108
Jones MC, Best PV, Catto GRD. Is nodular regenerative hyperplasia of the liver associated with azathioprine therapy after renal transplantation. Nephrol Dial Transplant 1988; 3: 330-3. (33 year old man developed minor elevations in liver tests starting 15 months after renal transplantation [bilirubin 1.0 mg/dL, AST 42 U/L, Alk P 185 U/L], later developing hepatomegaly and ascites; biopsy showed nodular regenerative hyperplasia). 3140109
Lemley DE, Delacy LM, Seeff LB, Ishak KG, Nashel DJ. Azathioprine induced hepatic veno-occlusive disease in rheumatoid arthritis. Ann Rheum Dis 1989; 48: 342-6. (59 year old man with rheumatoid arthritis developed abdominal pain 3 months after starting azathioprine with bilirubin 0.2 mg/dL, with minimal elevations in ALT and Alk P; azathioprine was continued and signs of portal hypertension arose 4 months later, biopsy showing sinusoidal obstruction syndrome). 2712618
Small P, Lichter M. Probable azathioprine hepatotoxicity: a case report. Ann Allergy 1989; 62: 518-20. (57 year old woman with rheumatoid arthritis and polymyositis developed AST and Alk P elevations 3 weeks after starting azathioprine, resolving with stopping and recurring with rechallenge, biopsies showed minimal nonspecific changes). 2735558
Ramalho HJ, Terra EG, Cartapatti E, Barberato JB, Alves VA, Gayotto LC, Abbud-Filho M. Hepatotoxicity of azathioprine in renal transplant recipients. Transplant Proc 1989; 21 (1 Pt 2): 1716-7. (2 women and 2 men, ages 28-49 years, developed cholestasis 2-18 months after renal transplant while on azathioprine [bilirubin 9.3-44 mg/dL, ALT 62-842 U/L, Alk P 1-3 times ULN], improving on stopping and reappearing within weeks on restarting azathioprine). 2652562
Tolman KG. Hepatotoxicity of antirheumatic drugs. J Rheumatol Suppl 1990; 22: 6-11. (Review of hepatotoxicity of drugs used in rheumatology; mentioning acute mixed hepatocellular-cholestatic injury from azathioprine). 2192059
Jeurissen ME, Boerbooms AM, van de Putte LB, Kruijsen MW. Azathioprine induced fever, chills, rash, and hepatotoxicity in rheumatoid arthritis. Ann Rheum Dis 1990; 49: 25-7. (Among 25 patients with rheumatoid arthritis, 3 developed fever and rash within 2 weeks of starting azathioprine; one had cholestasis [bilirubin 1.6 mg/dL, ALT 150 U/L, Alk P 810 U/L], resolving slowly after stopping and fever recurring upon rechallenge). 2138007
Singh G, Fries JF, Williams CA, Zatarain E, Spitz P, Bloch DA. Toxicity profiles of disease modifying antirheumatic drugs in rheumatoid arthritis. J Rheumatol 1991; 18: 188-94. (Analysis of side effects of 7 agents from the ARAMIS database including 2,479 patients [153 on azathioprine] with rheumatoid arthritis reported 5 instances of liver abnormalities, but no jaundice during ~228 patient years of exposure to azathioprine). 1673721
Horsmans Y, Rahier J, Geubel AP. Reversible cholestasis with bile duct injury following azathioprine therapy. A case report. Liver 1991; 11: 89-93. (67 year old man with polymyositis developed jaundice 3 months after starting azathioprine [bilirubin ~5.0 mg/dL, ALT ~120 U/L, Alk P 550 U/L], liver biopsy showing intrahepatic cholestasis and bile duct injury; resolving within 2 months of stopping). 2051906
Sterneck M, Wiesner R, Ascher N, Roberts J, Ferrell L, Ludwig J, Lake J. Azathioprine hepatotoxicity after liver transplantation. Hepatology 1991; 14: 806-10. (Two patients [58 year old woman and 41 year old man] developed jaundice 2 and 8 weeks after liver transplantation [bilirubin 33.8 and 7.1 mg/dL, AST 456 and 2965 U/L, Alk P not given and 349 U/L], liver biopsies showing centrilobular congestion, sinusoidal dilation and hemorrhagic necrosis suggesting vascular outflow obstruction, both improved on stopping azathioprine, one worsened on rechallenge). 1937385
Mion F, Napoleon B, Berger F, Chevallier M, Bonvoisin S, Descos L. Azathioprine induced liver disease: nodular regenerative hyperplasia of the liver and perivenous fibrosis in a patient treated for multiple sclerosis. Gut 1991; 32: 715-7. (37 year old man with multiple sclerosis developed variceal hemorrhage 7 years after starting azathioprine [100-150 mg/day], with biopsy showing nodular regeneration and perivascular fibrosis without inflammation). 2060883
Wagoner LE, Olsen SL, Bristow MR, O'Connell JB, Taylor DO, Lappe DL, Renlund DG. Cyclophosphamide as an alternative to azathioprine in cardiac transplant recipients with suspected azathioprine-induced hepatotoxicity. Transplantation 1993; 56: 1415-8. (29 of 320 cardiac transplant patients developed elevated liver enzymes on azathioprine, which improved when they were switched to cyclophosphamide 30-2014 days after transplant [mean bilirubin fell from 4.3 to 1.8 mg/dL, ALT 84 to 44 U/L, Alk P 184 to 149 U/L]; no rejection and all except one patient tolerated cyclophosphamide long term). 8279012
Gane E, Portmann B, Saxena R, Wong P, Ramage J, Williams R. Nodular regenerative hyperplasia of the liver graft after liver transplantation. Hepatology. 1994; 20: 88-94. (Nine cases of biopsy proven nodular regenerative hyperplasia in liver transplant recipients arising after 0.5-12 years; 6 presenting with ascites or varices and 3 without symptoms [bilirubin 0.5-5.1 mg/dL, AST 36-192 U/L, Alk P 159-1182 U/L], 5 improving on stopping azathioprine and 4 developing progressive hepatic failure; several had earlier biopsies showing venous outflow obstruction). 8020909
Dhillon AP, Burroughs AK, Hudson M, Shah N, Rolles K, Scheuer PJ. Hepatic venular stenosis after orthotopic liver transplantation. Hepatology 1994; 19: 106-11. (Retrospective review of 49 liver biopsies taken after liver transplantation identified 7 patients with venous outflow obstruction usually within 30 days of transplant, associated with endothelitis, only 5 on azathioprine suggesting that changes were due to rejection rather than drug). 8276346
Stetter M, Schmidl M, Krapf R. Azathioprine hypersensitivity mimicking Goodpasture's syndrome. Am J Kidney Dis 1994; 23: 874-7. PMID: PubMed Citation (Patient with renal transplant developed fever, arthralgias, diarrhea and pulmonary infiltrates within 7 days of starting azathioprine on three occasions, but later tolerated mercaptopurine suggesting hypersensitivity to nitroimidazole component of azathioprine). 8203372
Gross R. Hepatotoxicity of 6-mercaptopurine and azathioprine. Mayo Clin Proc 1994; 69: 498. (Letter in response to a review by Stark and Tremaine on use of thiopurines to treat Crohn disease mentioning the problem of hepatotoxicity of mercaptopurine and importance of monitoring for liver test abnormalities). 8170206
Laidlaw ST, Reilly JT, Suvarna SK. Fatal hepatotoxicity associated with 6-mercaptopurine therapy. Postgrad Med J 1995; 71: 639. (68 year old man developed jaundice [bilirubin 9.1 mg/dL, ALT 149 U/L, Alk P 143 U/L] after 5th cycle of chemotherapy for leukemia including mercaptopurine with progressive hepatic failure and death). 8545299
Kowdley KV, Keeffe EB. Hepatotoxicity of transplant immunosuppressive agents. Gastroenterol Clin North Am 1995; 24: 991-1001. (Review of hepatotoxicity of agents used in solid organ transplantation including azathioprine, which causes a broad range of hepatic injuries including transient ALT elevations, cholestasis, sinusoidal dilatation, veno-occlusive disease, peliosis and nodular regenerative hyperplasia with portal hypertension). 8749908
Knowles SR, Gupta AK, Shear NH, Sauder D. Azathioprine hypersensitivity-like reactions - a case report and a review of the literature. Clin Exp Dermatol 1995; 20: 353-6. (17 year old girl with vasculitis developed fever and leukopenia 15 days after starting azathioprine, with recurrence of fever within 24 hours of restarting; liver tests were normal). 8549000
Aguilar HI, Burgart LJ, Geller A, Rakela J. Azathioprine-induced lymphoma manifesting as fulminant hepatic failure. Mayo Clin Proc 1997; 72: 643-5. (50 year old woman with 15 year history of rheumatoid arthritis taking azathioprine for 5 years presented with jaundice [bilirubin 8.2 rising to 21.3 mg/dL, AST 185 to 1150 U/L, Alk P 600 to 810 U/L] resembling acute liver failure, biopsy showing hepatic involvement with T cell lymphoma). 9212766
Romagnuolo J, Sadowski DC, Lalor E, Jewell L, Thomson AB. Cholestatic hepatocellular injury with azathioprine: a case report and review of the mechanisms of hepatotoxicity. Can J Gastroenterol 1998; 12: 479-83. (63 year old man with Crohn's disease developed jaundice 9 weeks after starting azathioprine [bilirubin 8.0 mg/dL, AST 65 U/L, Alk P 896 U/L], liver biopsy showed intrahepatic cholestasis, resolved with stopping). 9812167
Griger DR, Higgs JB, Roane DW. Azathioprine hepatotoxicity is uncommon in patients with rheumatic diseases. J Clin Rheumatol 1999; 5: 60-4. (Retrospective review of 56 patients with rheumatic diseases treated with azathioprine, 41% had at least transient elevation in Alk P [146-302 U/L] or AST [39-234 U/L], but 80-90% fell to normal despite continuation and none were "clinically significant"). 19078358
Saeian K, Franco J, Komorowski RA, Adams MB. Hepatocellular carcinoma after renal transplantation in the absence of cirrhosis or viral hepatitis: a case series. Liver Transpl Surg 1999; 5: 46-9. (Two patients, ages 57 and 66 years, both men with renal transplant for 13 and 24 years, on prednisone and azathioprine, presented with HCC, but without cirrhosis or chronic hepatitis in the non-tumorous liver). 9873092
Mahadevan U, Tremaine WJ, Johnson T, Pike MG, Mays DC, Lipsky JJ, Sandborn WJ. Intravenous azathioprine in severe ulcerative colitis: a pilot study. Am J Gastroenterol 2000; 95: 3463-8. (9 hospitalized patients with refractory ulcerative colitis received 36 hour infusions of azathioprine; 5 had a clinical response and only one had hepatotoxicity [bilirubin not given, ALT 695 U/L, Alk P 474 U/L], resolving in 1 week). 11151878
Mok MY, Ng WL, Yuen MF, Wong RW, Lau CS. Safety of disease modifying anti-rheumatic agents in rheumatoid arthritis patients with chronic viral hepatitis. Clin Exp Rheumatol 2000; 18: 363-8. (Retrospective review of 29 Chinese patients with rheumatoid arthritis and chronic hepatitis B [n=23] or C [n=6] receiving disease modifying agents; one patient on azathioprine for 2.7 years developed reactivation of hepatitis B). 10895374
Cattan S, Wendum D, Chazouilleres O, Schmitz J, Gendre JP. Hepatocellular carcinoma and focal hepatic glycogenosis after prolonged azathioprine therapy. Hum Pathol 2000; 31: 874-6. (22 year old woman with 13 year history of Crohn disease and azathioprine therapy for 6 years developed HCC with focal hepatic glycogenosis in non-tumorous liver). 10923928
Evans WE, Hon YY, Bomgaars L, Coutre S, Holdsworth M, Janco R, Kalwinsky D, et al. Preponderance of thiopurine S-methyltransferase deficiency and heterozygosity among patients intolerant to mercaptopurine or azathioprine. J Clin Oncol 2001; 19: 2293-301. (Thiopurine S methyltransferase [TPMT] activity was low or deficient in 71% of patients with azathioprine hematologic toxicity, but among 6 patients with hepatoxicity none were deficient, 3 had intermediate and 3 normal levels of TPMT activity). 11304783
Russmann S, Zimmermann A, Krähenbühl S, Kern B, Reichen J. Veno-occlusive disease, nodular regenerative hyperplasia and hepatocellular carcinoma after azathioprine treatment in a patient with ulcerative colitis. Eur J Gastroenterol Hepatol 2001; 13: 287-90. (66 year old man with 12 year history of ulcerative colitis and 2 years of azathioprine therapy presented with jaundice, liver biopsy showing sinusoidal obstruction syndrome, nodular regenerative hyperplasia and HCC). 11293451
Schwab M, Schaeffeler E, Marx C, Fischer C, Lang T, Behrens C, Gregor M, et al. Azathioprine therapy and adverse drug reactions in patients with inflammatory bowel disease: impact of thiopurine S-methyltransferase polymorphism. Pharmacogenetics 2002; 12: 429-36. (Among 93 adults treated with azathioprine, thiopurine S-methyl transferase [TPMT] activities were normal in those with gastrointestinal [n=9] and liver toxicities [n=3], but were low in those with hematological toxicities). 12172211
Dubinsky MC, Vasiliauskas EA, Singh H, Abreu MT, Papadakis KA, Tran T, Martin P, et al. 6-thioguanine can cause serious liver injury in inflammatory bowel disease patients. Gastroenterology 2003; 125: 298-303. (Among 111 patients with inflammatory bowel disease treated with thioguanine at one institution, 27 [25%] developed abnormal liver tests [ALT 18-139 U/L; Alk P 35-221 U/L], correlating with higher methyl-metabolites of mercaptopurine and fall in platelet count [from 300,000 to 166,000], nodular regeneration found in 76% of 17 patients biopsied with abnormal liver tests, and 33% of nine with normal tests). 12891528
Sinico RA, Sabadini E, Borlandelli S, Cosci P, Di Toma L, Imbasciati E. Azathioprine hypersensitivity: report of two cases and review of the literature. J Nephrol 2003; 16: 272-6. (Two patients with systemic vasculitis developed fever, rash and malaise 10 and 20 days after starting azathioprine with prompt improvement on stopping and rapid relapse on restarting; no mention of liver test results as being abnormal). 12768076
Navarro JT, Ribera JM, Mate JL, Granada I, Juncà J, Batlle M, Millá F, et al. Hepatosplenic T-gammadelta lymphoma in a patient with Crohn's disease treated with azathioprine. Leuk Lymphoma. 2003; 44: 531-3. (35 year old man with 15 year history of Crohn disease and 5 year history of azathioprine therapy presented with fever, hepatomegaly and HSTCL). 12688327
de Abajo FJ, Montero D, Madurga M, GarciaRodriguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Analysis of UK General Practice Research Database found 128 cases of suspected drug induced liver injury [2.4 per 100,000 person-years], 2 anicteric cases were attributed to azathioprine, yielding an odds ratio of 10.5). 15206996
Kontorinis N, Agarwal K, Gondolesi G, Fiel MI, O'Rourke M, Schiano TD. Diagnosis of 6 mercaptopurine hepatotoxicity post liver transplantation utilizing metabolite assays. Am J Transplant 2004; 4: 1539-42. (Two women, ages 46 and 53 years, with liver transplants developed jaundice 5 and 3 months after starting mercaptopurine [bilirubin 11.7 and 8.0 mg/dL, ALT 108 and 392 U/L, Alk P 464 and 395 U/L], resolving within 1-2 months of stopping; neither had TPMT deficiency). 15307844
Nygaard U, Toft N, Schmiegelow K. Methylated metabolites of 6-mercaptopurine are associated with hepatotoxicity. Clin Pharmacol Ther 2004; 75: 274-81. (High frequency of ALT elevations occurred in children with acute leukemia treated with mercaptopurine usually resolving with stopping or lowering the dose; ALT elevations were associated with higher doses and higher levels of methylated metabolites of mercaptopurine). 15060506
Reuther LO, Vainer B, Sonne J, Larsen NE. Thiopurine methyltransferase(TPMT) genotype distribution in azathioprine-tolerant and -intolerant patients with various disorders. The impact of TPMT genotyping in predicting toxicity. Eur J Clin Pharmacol 2004; 59: 797-801. (Weak correlation found between azathioprine intolerance and TPMT mutations). 14634700
de Boer NK, Mulder CJ, van Bodegraven AA. Myelotoxicity and hepatotoxicity during azathioprine therapy. Neth J Med 2005; 63: 444-6. (38 year old man with Crohn's disease was found to have abnormal liver tests and portal hypertension 3 years after starting azathioprine [bilirubin 2.1 mg/dL, ALT 53 U/L, Alk P 141 U/L], improving upon stopping). 16397313
Heckmann JM, Lambson EM, Little F, Owen EP. Thiopurine methyltransferase(TPMT) heterozygosity and enzyme activity as predictive tests for the development of azathioprine-related adverse events. J Neurol Sci 2005; 231: 71-80. (7 of 129 neurological patients on azathioprine developed hepatotoxicity; testing for TPMT activity or mutations had low predictive value). 15792824
Sparrow MP, Hande SA, Friedman S, Lim WC, Reddy SI, Cao D, Hanauer SB. Allopurinol safely and effectively optimizes thioguanine metabolites in inflammatory bowel disease patients not responding to azathioprine and mercaptopurine. Aliment Pharmacol Ther 2005; 22: 441-6. (Adding allopurinol to azathioprine therapy led to higher thioguanine and methyl-mercaptopurine levels, thus allowing for reduction in azathioprine dose, and theoretically better efficacy, lower toxicity). 16128682
Daniel F, Cadranel JF, Seksik P, Cazier A, Duong Van Huyen JP, Ziol M, Coutarel P, et al. Azathioprine induced nodular regenerative hyperplasia in IBD patients. Gastroenterol Clin Biol 2005; 29: 600-34. (Four men, ages 26 to 46 years, with inflammatory bowel disease developed nodular regenerative hyperplasia 6-12 months after starting azathioprine, presenting with liver test abnormalities and decrease in platelet counts, improving with stopping including slight increase in platelet count: Azathioprine Case 3). 15980758
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Among 446 cases of drug induced liver injury collected in Spain between 1984-2004, azathioprine accounted for 6 cases, ranking 14th; injury usually cholestatic, no fatalities). 16083708
Seiderer J, Zech CJ, Diebold J, Schoenberg SO, Brand S, Tillack C, Göke B, Ochsenkühn T. Nodular regenerative hyperplasia: a reversible entity associated with azathioprine therapy. Eur J Gastroenterol Hepatol 2006; 18: 553-5. (54 year old developed jaundice 5 months after starting azathioprine for Crohn's disease [bilirubin 7.5 mg/dL, but normal serum enzymes], biopsy showing nodular regenerative hyperplasia, improvement on stopping). 16607155
Chen SC, Cummings OW, Hartley MP, Filomena CA, Cho WK. Hepatocellular carcinoma occurring in a patient with Crohn's disease treated with both azathioprine and infliximab. Dig Dis Sci 2006; 51: 952-5. (28 year old woman with 14 year history of Crohn disease on azathioprine and infliximab was found to have 2 cm liver mass on routine imaging of the liver, biopsy showing focal hepatic glycogenosis). 16670938
Heneghan MA, Allan ML, Bornstein JD, Muir AJ, Tendler DA. Utility of thiopurine methyltransferase genotyping and phenotyping, and measurement of azathioprine metabolites in the management of patients with autoimmune hepatitis. J Hepatol 2006; 45: 584-91. (Among 86 patients with autoimmune hepatitis treated with azathioprine, TPMT mutations did not predict toxicities, one patient developed hepatotoxicity with rise in ALT to 3 times ULN that improved with dose reduction). 16876902
Shaye OA, Yadegari M, Abreu MT, Poordad F, Simon K, Martin P, Papadakis KA, et al. Hepatotoxicity of 6-mercaptopurine (6-MP) and azathioprine (AZA) in adult IBD patients. Am J Gastroenterol 2007; 102: 2488-94. (Among 173 adult patients with inflammatory bowel disease treated with azathioprine or mercaptopurine, 8 developed ALT elevations greater than twice ULN [bilirubin 0.3-2.4 mg/dL, ALT 58-434 U/L, Alk P 54-130 U/L], resolving with stopping or lowering dose; toxicity had weak association with higher methyl metabolites in serum). 17764490
Gisbert JP, Luna M, González-Lama Y, Pousa ID, Velasco M, Moreno-Otero R, Maté J. Liver injury in inflammatory bowel disease: long-term follow-up study of 786 patients. Inflamm Bowel Dis 2007; 13: 1106-14. (Long term follow up of 138 patients treated with azathioprine or mercaptopurine; incidence of any abnormal liver test was 7.1% per year, values >twice ULN occurred in only 2.6% and often resolved spontaneously; 5 of 49 required discontinuation). 17455203
Contreras AM, Monteón FJ, Flores MR, Mendoza-Sánchez F, Ruiz I. Drug-related hepatotoxicity in a renal transplant recipient with long-term survival and hepatitis C. Ann Hepatol 2007; 6: 70-3. (53 year old man with renal transplant developed ALT elevations during long term azathioprine therapy, but was subsequently found to have acquired chronic hepatitis C as a possible reason for the liver injury). 17297434
Samarasena J, Borgaonkar M. Development of hepatocellular carcinoma in a patient with Crohn's disease treated with azathioprine. Dig Dis Sci 2007; 52: 2748-50. (37 year old man with 18 year history of Crohn disease and 2 years of azathioprine therapy, presented with abdominal pain and an unresectable HCC [bilirubin 1.0, ALT 23 U/L, Alk P 163 U/L], but no radiologic or clinical evidence of cirrhosis). 17404860
Lees CW, Maan AK, Hansoti B, Satsangi J, Arnott DR. Tolerability and safety of mercaptopurine in azathioprine-intolerant patients with inflammatory bowel disease. Aliment Pharmacol Ther 2008; 27: 220-7. (Retrospective analysis of 61 patients with inflammatory bowel disease who were intolerant to azathioprine; 36 [59%] were able to tolerate mercaptopurine including 3 of 9 with hepatotoxicity). 17988235
Ehmsen L, Marko C, Breidert M. [Portal vein hypertension during azathioprine therapy in patients with Crohn's disease - a frequent phenomenon?]. Dtsch Med Wochenschr 2008; 133: 950-3. German. PMID: 18431703 (45 year old man with Crohn's disease on azathioprine for 4 years developed variceal hemorrhage [bilirubin 4.1 mg/dL, normal ALT, platelets 84,000/μL] and was found to have nodular regenerative hyperplasia on liver biopsy and subsequently improved on stopping azathioprine).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 were attributed to mercaptopurine, but none to azathioprine or thioguanine). 18955056
Rahhal RM, Bishop WP. Initial clinical experience with allopurinol-thiopurine combination therapy in pediatric inflammatory bowel disease. Inflamm Bowel Dis 2008; 14: 1678-82. (13 patients were treated with allopurinol and dose reduction of azathioprine [by ~60%] with overall increase in 6-thioguanine and decrease in methyl-metabolites; ALT elevations improved in all). 18521913
Ansari A, Elliott T, Baburajan B, Mayhead P, O'Donohue J, Chocair P, Sanderson J, Duley J. Long-term outcome of using allopurinol co-therapy as a strategy for overcoming thiopurine hepatotoxicity in treating inflammatory bowel disease. Aliment Pharmacol Ther 2008; 28: 734-41. (11 patients with inflammatory bowel disease who developed hepatotoxicity within 1-8 weeks of starting azathioprine [n=10] or mercaptopurine [n=1] were treated with allopurinol and low doses of the thiopurine; 9 tolerated long term therapy without recurrence). 19145729
Xin HW, Xiong H, Wu XC, Li Q, Xiong L, Yu AR. Relationships between thiopurine S-methyltransferase polymorphism and azathioprine-related adverse drug reactions in Chinese renal transplant recipients. Eur J Clin Pharmacol 2009; 65: 249-55. (Association found between TPMP activity and hemato- but not hepatotoxicity; only 2 of 16 patients with hepatotoxicity were heterozygous for TPMT mutations, none were homozygous). 19048245
Hindorf U, Johansson M, Eriksson A, Kvifors E, Almer SH. Mercaptopurine treatment should be considered in azathioprine intolerant patients with inflammatory bowel disease. Aliment Pharmacol Ther 2009; 29: 654-61. (Analysis of usefulness of measuring thiopurine metabolites in management of 238 patients with autoimmune hepatitis on azathioprine, finding it useful only in managing patients with a poor response; patients with hepatotoxicity were not able to tolerate switch to mercaptopurine). 19183142
Murakami A, Tanaka Y, Ueda M, Nagano Y, Kunisaki R, Morimoto M, Enaka M, et al. Hepatocellular carcinoma occurring in a young Crohn's disease patient. Pathol Int 2009; 59: 492-6. (25 year old man with 12 year history of Crohn disease presented with hepatocellular carcinoma approximately one year after starting infliximab; no other risk factors identified; review of literature identified 7 cases in patients with Crohn's, mean age 20 years, all had received azathioprine and two infliximab). 19563414
Takatsu N, Matsui T, Murakami Y, Ishihara H, Hisabe T, Nagahama T, Maki S, et al. Adverse reactions to azathioprine cannot be predicted by thiopurine S-methyltransferase genotype in Japanese patients with inflammatory bowel disease. J Gastroenterol Hepatol 2009; 24: 1258-64. (TPMT deficiency variants were rare [~2%] in Japanese and were not increased among those with azathioprine intolerance due to toxicity; 2 cases had hepatotoxicity). 19682195
Germani G, Pleguezuelo M, Villamil F, Vaghjiani S, Tsochatzis E, Andreana L, Burroughs AK. Azathioprine in liver transplantation: a reevaluation of its use and a comparison with mycophenolate mofetil. Am J Transplant 2009; 9: 1725-31. (Review of literature suggests that there is no evidence for added benefit of mycophenolate over azathioprine for prevention of rejection or graft survival after liver transplantation; no discussion of hepatotoxicity). 19538488
Roda G, Caponi A, Belluzzi A, Roda E. Severe cholestatic acute hepatitis following azathioprine therapy in a patient with ulcerative pancolitis. Dig Liver Dis 2009; 41: 914-5. (50 year old man with ulcerative colitis developed jaundice 20 days after starting azathioprine [50 mg daily] [bilirubin 14.8 rising to 26.8 mg/dL, ALT 225 U/L, Alk P 952 U/L], with jaundice lasting 3 months but ultimately complete recovery). 19376754
Moran G, Dillon J, Green J. Crohn's disease, hepatosplenic T-cell lymphoma and no biological therapy: are we barking up the wrong tree? Inflamm Bowel Dis 2009; 15: 1281-2. (Although fewer than 200 cases of hepatosplenic T cell lymphoma [HSTCL] have been described in the literature, 23 have occurred in patients with inflammatory bowel disease, all of whom were on thiopurines and 16 also on anti-tumor necrosis factor antagonists [anti-TNF]; the authors describe a 23 year old man with ulcerative colitis treated with azathioprine for 7 years without anti-TNF who developed HSTCL). 19067412
Beigel F, Jürgens M, Tillack C, Subklewe M, Mayr D, Göke B, Brand S, et al. Hepatosplenic T-cell lymphoma in a patient with Crohn's disease. Nat Rev Gastroenterol Hepatol 2009; 6: 433-6. (58 year old man with 35 year history of Crohn disease on azathioprine for 5 years developed HSTCL). 19575026
Murakami A, Tanaka Y, Ueda M, Nagano Y, Kunisaki R, Morimoto M, Enaka M, et al. Hepatocellular carcinoma occurring in a young Crohn's disease patient. Pathol Int 2009; 59: 492-6. (25 year old Japanese man with 12 year history of Crohn disease on azathioprine and infliximab presented with abdominal pain and 8 cm HCC without cirrhosis in the non-tumorous liver). 19563414
Miura H, Kawaguchi T, Takazoe M, Kitamura S, Yamada H. Hepatocellular carcinoma and Crohn's disease: a case report and review. Intern Med 2009; 48: 815-9. (52 year old Japanese man with 36 year history of Crohn disease, but never treated with thiopurines presented with hepatic mass, found to be HCC with chronic hepatitis in non-tumorous liver tissue). 19443977
Thai A, Prindiville T. Hepatosplenic T-cell lymphoma and inflammatory bowel disease. J Crohns Colitis 2010; 4: 511-22. (Review of the association of HSTCL and inflammatory bowel disease). 21122554
Ishida M, Naka S, Shiomi H, Tsujikawa T, Andoh A, Nakahara T, Saito Y, et al. Hepatocellular carcinoma occurring in a Crohn's disease patient. World J Gastroenterol 2010; 16: 3215-8. (37 year old Japanese man with 7 year history of Crohn disease developed 3 to 4 cm HCC, with focal hepatic glycogenosis without cirrhosis in the non-tumorous liver and with successful resection). 20593510
Ochenrider MG, Patterson DJ, Aboulafia DM. Hepatosplenic T-cell lymphoma in a young man with Crohn's disease: case report and literature review. Clin Lymphoma Myeloma Leuk 2010; 10: 144-8. (18 year old man with 5 year history of Crohn disease treated with mercaptopurine developed HSTCL [bilirubin and ALT levels normal]). 20371449
Ben Salem C, Ben Salah L, Belajouza C, Bouraoui K. Azathioprine-induced severe cholestatic hepatitis in patient carrying TPMT*3C polymorphism. Pharm World Sci 2010; 32: 701-3. (40 year old with pemphigus foliaceus developed jaundice 3 weeks after starting azathioprine [bilirubin 24.2 mg/dL, ALT 1140 U/L, Alk P 301 U/L], with resolution within months of stopping). 20972624
Bermejo F, López-Sanromán A, Algaba A, Van-Domselaar M, Gisbert JP, García-Garzón S, Garrido E, et al. Mercaptopurine rescue after azathioprine-induced liver injury in inflammatory bowel disease. Aliment Pharmacol Ther 2010; 31: 120-4. (Retrospective analysis of 31 patients with inflammatory bowel disease who were switched from azathioprine to mercaptopurine because of liver toxicity; in 87%, mercaptopurine was tolerated without evidence of further toxicity). 19709096
Hunt CM. Mitochondrial and immunoallergic injury increase risk of positive drug rechallenge after drug-induced liver injury: a systematic review. Hepatology 2010; 52: 2216-22. (Systematic review of literature on drug rechallenge after acute injury; positive rechallenge after azathioprine hepatotoxicity is common and can be severe). 21105110
Andrejic J, Rojas-Balcazar J, Dennis M, Berkelhammer C. Azathioprine-induced hypersensitivity hepatitis: tolerance to 6-mercaptopurine. Inflamm Bowel Dis. 2010; 16: 1828-9. (50 year old man with ulcerative colitis developed jaundice 4 weeks after starting azathioprine [bilirubin 4.6 mg/dL, ALT 1077 U/L, Alk P 361 U/L], resolving upon stopping and not recurring when treated with mercaptopurine [for up to 6 years]). 20196148
Ishida M, Naka S, Shiomi H, Tsujikawa T, Andoh A, Nakahara T, Saito Y, et al. Hepatocellular carcinoma occurring in a Crohn's disease patient. World J Gastroenterol 2010; 16: 3215-8. (37 year old Japanese man treated with azathioprine for 8 years developed liver cancer without cirrhosis but with glycogenosis present; review of 10 reported cases, all without cirrhosis). 20593510
Bryant DL, Miles CJ, Gearry RB. Nodular regenerative hyperplasia of the liver secondary to azathioprine in a patient with inflammatory bowel disease. N Z Med J 2010; 123: 74-6. (54 year old man developed ascites and splenomegaly 18 months after starting azathioprine for Crohn disease, biopsy showing nodular regenerative hyperplasia, improving upon stopping). 20581898
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury of which none were attributed to azathioprine or other thiopurines). 20949552
Okan G, Vural P, Peker O, Colakoglu E, Saruc M. Azathioprine-induced liver injury in a patient with multiple autoimmune syndrome. J Dermatolog Treat 2010; 21: 357-60. (39 year old man with autoimmune disease developed abnormal liver tests 3 weeks after starting azathioprine [bilirubin normal, GGT 2768 U/L, Alk P 306 U/L], resolving within 2 months of stopping). 20443662
López-Martín C, de la Fuente-Fernández E, Corbatón P, Sánchez MC, Gisbert JP. [Nodular regenerative hyperplasia: azathioprine-induced hepatotoxicity in a patient with Crohn's disease]. Gastroenterol Hepatol 2011; 34: 16-9. Spanish. PMID: 21168244 (53 year old man developed abnormal liver tests after 5 years of azathioprine therapy [7 months after dose increase] for Crohn disease [bilirubin 2.2 mg/dL, ALT 61 U/L, Alk P 284 U/L], with esophageal varices and biopsy showing nodular regenerative hyperplasia; slow improvement upon stopping).
Blogowski W, Marlicz W, Smereczynski A, Lawniczak M, Lewosiuk A, Starzynska T. Nodular regenerative liver hyperplasia as a complication of azathioprine-containing immunosuppressive treatment for Crohn's disease. Immunopharmacol Immunotoxicol 2011; 33: 398-402. (40 year old woman with Crohn disease developed nodular regenerative hyperplasia [splenomegaly and varices] 3 years after starting azathioprine). 20726808
Seksik P, Mary JY, Beaugerie L, Lémann M, Colombel JF, Vernier-Massouille G, Cosnes J. Incidence of nodular regenerative hyperplasia in inflammatory bowel disease patients treated with azathioprine. Inflamm Bowel Dis 2011; 17: 565-72. (Among 1888 patients with inflammatory bowel disease treated with azathioprine for median of 2.5 years, 15 developed nodular regenerative hyperplasia, 0.6% at 5 and 1.3% at 10 years; predictive factors were male gender and history of small bowel resection). 20848502
Wree A, Dechêne A, Herzer K, Hilgard P, Syn WK, Gerken G, Canbay A. Steroid and ursodeoxycholic Acid combination therapy in severe drug-induced liver injury. Digestion 2011; 84: 54-9. (15 patients with various forms of drug induced liver injury were treated with ursodiol [750-1500 mg/day] and prednisone [various regimens] for 4-10 weeks; all patients improved and rate of improvement was faster than in a historical control group). 21304237
Aithal GP. Hepatotoxicity related to antirheumatic drugs. Nat Rev Rheumatol 2011; 7: 139-50. (Review of the hepatotoxicity of antirheumatic drugs including azathioprine; acute cholestatic injury occurs in 1:1000 treated subjects, mechanism may be immunologic, metabolic, and/or genetic). 21263458
Meggitt SJ, Anstey AV, Mohd Mustapa MF, Reynolds NJ, Wakelin S. British Association of Dermatologists' guidelines for the safe and effective prescribing of azathioprine 2011. Br J Dermatol 2011; 165: 711-34. (Guidelines for the use of azathioprine in skin diseases including systemic lupus, dermatomyositis and pemphigus, mentions that mild liver enzyme changes are "not uncommon" and may not require alteration of therapy, while severe hepatotoxicity is rare but does). 21950502
Adam de Beaumais T, Fakhoury M, Medard Y, Azougagh S, Zhang D, Yakouben K, Jacqz-Aigrain E. Determinants of mercaptopurine toxicity in paediatric acute lymphoblastic leukemia maintenance therapy. Br J Clin Pharmacol 2011;71: 575-84. (66 children with acute leukemia treated with mercaptopurine were tested for thiopurine methyltransferase [TPMT] and inosine pyrophosphatase (ITPA) polymorphisms and for serum levels of mercaptopurine and metabolites; those with higher levels of methyl metabolites [which varied by ITPA genotype] were more likely to have hepatotoxicity, present in 84% of participants). 21395650
Calabrese E, Hanauer SB. Assessment of non-cirrhotic portal hypertension associated with thiopurine therapy in inflammatory bowel disease. J Crohns Colitis 2011; 5: 48-53. (Review of thiopurine toxicity and its management, highlighting a case of nodular regenerative hyperplasia in a patient with Crohn's colitis treated with mercaptopurine). 21272804
Srirajaskanthan R, Valliani D. Azathioprine induced hepatitis in patients with inflammatory bowel disease. Int J Clin Pharm 2011; 33: 724-5. (Two patients developed symptoms, jaundice and ALT elevations on azathioprine therapy, both having normal TPMT levels; few details given). 21892694
Rashidi A, Lee ME, Fisher SI. Hepatosplenic αβ T-cell lymphoma associated with azathioprine therapy. Int J Hematol 2012; 95: 592-4. (47 year old woman with systemic lupus erythematosus on long term azathioprine, rituximab and prednisone developed HSTCL). 22527855
Choudhary NS, Gupta S, Chawla YK, Duseja A, Dhiman RK, Das A. Azathioprine induced liver injury: a case report. Dig Dis Sci 2012; 57: 1717-8. (61 year old man developed jaundice 16 days after starting azathioprine [bilirubin 9.2 rising to 21.6 mg/dL, ALT 138 U/L, Alk P 3 times ULN], resolving within 6 months of stopping). 22526581
van Asseldonk DP, Seinen ML, de Boer NK, van Bodegraven AA, Mulder CJ. Hepatotoxicity associated with 6-methyl mercaptopurine formation during azathioprine and 6-mercaptopurine therapy does not occur on the short-term during 6-thioguanine therapy in IBD treatment. J Crohns Colitis 2012; 6: 95-101. (Among 19 patients with inflammatory bowel disease who developed serum enzyme elevations during azathioprine or mercaptopurine therapy, none developed liver injury during thioguanine therapy and mean ALT values decreased [64 to 20 U/L]). 22261533
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 4 attributed to azathioprine for an estimated incidence of 1 per 133 treated subjects; all cases were symptomatic, but anicteric). 23419359
Hoentjen F, Seinen ML, Hanauer SB, de Boer NK, Rubin DT, Bouma G, Harrell LE, van Bodegraven AA. Safety and effectiveness of long-term allopurinol-thiopurine maintenance treatment in inflammatory bowel disease. Inflamm Bowel Dis 2013; 19: 363-9. (Among 36 patients with inflammatory bowel disease who developed ALT elevations during thiopurine therapy who were treated with allopurinol and low doses of thiopurines, ALT levels became normal in 24 and mean values decreased from 38 [range 21-84] to 21 [range 15-26] U/L). 22605661
Chun JY, Kang B, Lee YM, Lee SY, Kim MJ, Choe YH. Adverse events associated with azathioprine treatment in korean pediatric inflammatory bowel disease patients. Pediatr Gastroenterol Hepatol Nutr 2013; 16: 171-7. (Among 174 Korean children with inflammatory bowel disease treated with azathioprine between 2002 and 2012, 98 [56%] had an adverse event, including 5 [2.9%] with "hepatitis" arising after 1 to 30 months [mean ALT 140 U/L] and resolving spontaneously in all without dose reduction or even temporary discontinuation). 24224150
Patel VN, Kaelber DC. Using aggregated, de-identified electronic health record data for multivariate pharmacosurveillance: A case study of azathioprine. J Biomed Inform 2013 Oct 28. pii: S1532-0464(13)00161-5. (Analysis of electronic health records of 10 million persons identified 14,580 who received azathioprine, among whom 14% had an elevation in ALT, AST or bilirubin which was not significantly higher than rates of elevations with other antirheumatic agents). 24177317
Kennedy NA, Rhatigan E, Arnott ID, Noble CL, Shand AG, Satsangi J, Lees CW. A trial of mercaptopurine is a safe strategy in patients with inflammatory bowel disease intolerant to azathioprine: an observational study, systematic review and meta-analysis. Aliment Pharmacol Ther 2013; 38: 1255-66. (Retrospective study and systematic review of literature reports that 81% of persons who developed azathioprine hepatotoxicity were able to tolerate mercaptopurine). 24117596
Wieser V, Gerner R, Moschen AR, Tilg H. Liver complications in inflammatory bowel diseases. Dig Dis 2013; 31: 233-8. (Review of the hepatic manifestations of inflammatory bowel disease including drug induced liver injury from the thiopurines, antitumor necrosis factor agents and methotrexate). 24030232
Ruiz-Clavijo D, Arín A, Vila JJ, Albéniz E, Picazo R, Casi M. [Azathioprine-induced hepatotoxicity in a patient with Crohn's disease]. An Sist Sanit Navar 2013; 36: 353-6. Spanish. PMID: 24008542 (35 year old person with Crohn disease was found to have abnormal liver tests and esophageal varices 14 months after starting azathioprine [bilirubin and ALT normal, Alk P 248 U/L], improving upon stopping).
Chaparro M, Ordás I, Cabré E, Garcia-Sanchez V, Bastida G, Peñalva M, Gomollón F, et al. Safety of thiopurine therapy in inflammatory bowel disease: long-term follow-up study of 3931 patients. Inflamm Bowel Dis 2013; 19: 1404-10. (Among 3931 patients with inflammatory bowel disease who were treated with a thiopurine [95% with azathioprine] and were followed in a prospective Spanish nationwide database, 156 [4%] developed hepatotoxicity [ALT above 2 times ULN] of whom 88 [56%] stopped therapy, but only 2 of 23 [8%] who restarted, redeveloped liver toxicity). 23665964
Mazor Y, Koifman E, Elkin H, Chowers Y, Krivoy N, Karban A, Efrati E. Risk factors for serious adverse effects of thiopurines in patients with Crohn's disease. Curr Drug Saf 2013; 8: 181-5. (Among 176 patients with Crohn disease treated with mercaptopurine [n=131] or azathioprine [n=45], 24 developed a severe adverse event, risk factors being older age, smoking and the null genotype variant of GSTM1). 23845145
Appell ML, Wagner A, Hindorf U. A skewed thiopurine metabolism is a common clinical phenomenon that can be successfully managed with a combination of low-dose azathioprine and allopurinol. J Crohns Colitis 2013; 7: 510-3. (A 59 year old woman with Crohn disease developed ALT elevations [~160 U/L] 2 months after starting azathioprine [150 mg/day], which resolved on stopping and recurred on restarting [~200 U/L], with high levels of serum methylated metabolites and low levels of thioguanine nucleotide [TGN]; subsequent use of low doses of azathioprine [50 mg daily] and allopurinol was well tolerated and associated with correction of the serum metabolite pattern). 23168376
Dooremont D, Decaestecker J, De Wulf D, Ghillebert G, Van Vlierberghe H, Van Dorpe J, Baert F. Azathioprine induced serious portal hypertension: a case series of three IBD patients and review of the literature. Acta Gastroenterol Belg 2013; 76: 342-6. (Ordered). 24261031
León-Montañes R, Trigo-Salado C, Leo-Carnerero E, de-la-Cruz-Ramírez MD, Herrera-Justiniano JM, Márquez-Galán JL. Treatment with adalimumab in a patient with regenerative nodular hyperplasia secondary to azathioprine. Rev Esp Enferm Dig 2013; 105: 168-70. (47 year old man with Crohn disease developed evidence of liver injury one year after starting azathioprine [bilirubin 2.0 mg/dL, ALT 69 U/L, Alk P 207 U/L, platelets 120,000] with hepatosplenomegaly and biopsy showing nodular regenerative hyperplasia; was switched from azathioprine to adalimumab wtih no further worsening of liver condition). 23735025
Pallavicino F, Pellicano R, Reggiani S, Simondi D, Sguazzini C, Bonagura AG, Cisarò F, et al. Inflammatory bowel diseases and primary sclerosing cholangitis: hepatic and pancreatic side effects due to azathioprine. Eur Rev Med Pharmacol Sci 2013; 17: 84-7. (Among 43 patients with sclerosing cholangitis and inflammatory bowel disease followed at a referral center in Italy, 12 were treated with ursodiol and azathioprine of whom 4 developed "hepatic toxic reactions"; no details provided). 23329527
Selvaraj SA, Chairez E, Wilson LM, Lazarev M, Bass EB, Hutfless S. Use of case reports and the Adverse Event Reporting System in systematic reviews: overcoming barriers to assess the link between Crohn's disease medications and hepatosplenic T-cell lymphoma. Syst Rev 2013; 2: 53. (Review of the literature and spontaneous reports made to the FDA of HSTCL and medication use, identified 37 cases, ages 12 to 79 [mean 30] years; 86% male; disease duration 4 to 35 [mean 10] years; 96% having received thiopurines, 76% biologics; survival poor [8%]). 23826928
Bašić Kinda S, Duraković N, Dotlić S, Serventi Seiwerth R, Davidović Mrsić S, Dubravčić K, Aurer I. Hepatosplenic αβ T-cell lymphoma arising after long-term azathioprine therapy successfully treated with allogeneic bone marrow transplant. Leuk Lymphoma 2013; 54: 1334-5. (Report of a patient with Crohn disease who developed HSTCL after 7 years of azathioprine therapy, few details provided). 23083012
Björnsson ES. Epidemiology and risk factors for idiosyncratic drug-induced liver injury. Semin Liver Dis 2014; 34: 115-22. (Review of the epidemiology of drug induced liver injury mentions that the estimated crude risk of hepatotoxicity from azathioprine is 1 per 1,103 exposed patients). 24879977
Chertoff J, Alam S, Black M, Elgendy IY. Azathioprine-induced hepatitis and cholestasis occurring 1 year after treatment. BMJ Case Rep 2014; 2014. pii: bcr2014206859. (47 year old man with myasthenia gravis developed jaundice 1 year after starting azathioprine [200 mg daily] [bilirubin 16.1 mg/dL, ALT 102 U/L, Alk P not given], with resolution within 1 month of stopping). 25471111
Trabelsi AB, Hamami E, Souguir A, Ksiaa M, Ajmi S, Jmaa A. Suspected azathioprine induced liver cirrhosis: an unusual side effect. Pan Afr Med J 2014; 17: 174. (56 year old woman with long standing Crohn disease developed cirrhosis 4 years after starting azathioprine despite normal serum ALT levels, but few details provided). 25392720
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to azathioprine or mercaptopurine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 10 [1.3%] cases were attributed to azathioprine and 9 [1.2%] to mercaptopurine, thus representing the 13th and 14th most frequent prescription drugs implicated). 25754159
Botros Y, Mathews M, Patel H, Shah N, Baddoura W, de la Torre A. Recurrent hepatocellular carcinoma in patient with Crohn's disease: incidental or expected outcome of azathioprine? Case Rep Gastrointest Med 2015; 2015: 939136. (62 year old man with Crohn disease and azathioprine therapy for 21 years, developed HCC with recurrence after resection; no mention of cirrhosis). 26788381
Jack KL, Koopman WJ, Hulley D, Nicolle MW. A review of azathioprine-associated hepatotoxicity and myelosuppression in myasthenia gravis. J Clin Neuromuscul Dis 2016; 18: 12-20. (Among 571 patients with myasthenia gravis treated with azathioprine at a referral center in Canada, 87 [15%] developed hepatotoxicity [27 with concurrent myelotoxicity], mostly manifested by asymptomatic rise in GGT levels, but 31 [5%] with symptoms and 1 with cholestatic hepatitis). 27552384
Brinkert F, Arrenberg P, Krech T, Grabhorn E, Lohse A, Schramm C. Two cases of hepatosplenic T-cell lymphoma in adolescents treated for autoimmune hepatitis. Pediatrics 2016; 138. pii: e20154245. (Two patients who developed HSTCL during azathioprine therapy of autoimmune hepatitis: 21 year old man treated for 5 years and an 18 year old female treated for 4 years, both presenting with hepatosplenomegaly, fever and pancytopenia). 27516526
Suárez Ferrer C, Llop Herrera E, Calvo Moya M, Vera Mendoza MI, González Partida I, González Lama Y, Matallana Royo V, et al. Idiopathic portal hypertension regarding thiopurine treatment in patients with inflammatory bowel disease. Rev Esp Enferm Dig 2016; 108: 79-83. (Among 1419 patients with inflammatory bowel disease followed at a referral center in Spain, 927 were treated with thiopurines, of whom 63 [7%] developed liver injury, mostly hepatotoxicity that resolved with dose modification or discontinuation, but 4 had portal hypertension and probable nodular regenerative hyperplasia [ages 42 to 72 years, treated for 2.5-10 years, bilirubin 0.4-2.2 mg/dL, ALT 21-65 U/L, platelet counts 60,000-100,000]). 26838489
van de Meeberg MM, Derikx LA, Sinnige HA, Nooijen P, Schipper DL, Nissen LH. Hepatosplenic T-cell lymphoma in a 47-year-old Crohn's disease patient on thiopurine monotherapy. World J Gastroenterol 2016; 22: 10465-70. (47 year old man with Crohn disease on azathioprine therapy developed HSTCL, few details provided). 28058028
Heron V, Fortinsky KJ, Spiegle G, Hilzenrat N, Szilagyi A. Resected hepatocellular carcinoma in a patient with Crohn's disease on azathioprine. Case Rep Gastroenterol 2016; 10: 50-6. (61 year old woman with 30 year history of Crohn disease and 10 years of azathioprine therapy presented with liver mass with HCC on biopsy without cirrhosis, but no malignancy at time of resection several months later). 27403102
Björnsson ES, Gu J, Kleiner DE, Chalasani N, Hayashi PH, Hoofnagle JH; DILIN Investigators. Azathioprine and 6-mercaptopurine-induced liver injury: clinical features and outcomes. J Clin Gastroenterol 2017; 51: 63-9. (Among 12 cases of azathioprine induced liver injury enrolled in a prospective US database, all patients were adults being treated for autoimmune conditions; latency ranged from 3 days to more than a year, but usually was within 3 months of starting or a major dose escalation, the disease being anicteric in 4, icteric in 8, severe in 2, with initial bilirubin 0.6-31.8 [mean=6.7] mg/dL, ALT 116-625 [mean=254] U/L, Alk P 77-412 [mean=190] U/L, and liver biopsy showing cholestatic hepatitis and mild-to-moderate bile duct injury but no duct loss; cases due to mercaptopurine [n=10] tended to be similar in clinical characteristics, although somewhat more severe). 27648552
Siramolpiwat S, Sakonlaya D. Clinical and histologic features of azathioprine-induced hepatotoxicity. Scand J Gastroenterol. 2017;52:876-880.. (Among 293 patients treated with azathioprine at a single medical center in Thailand between 2010 and 2015, 8 [2.7%] developed evidence of hepatotoxicity with a mean latency of 86 days [range 7 to 236], with peak median ALT 295 U/L, Alk P 167 U/L, bilirubin 1.0 mg/dL; 4 with symptoms, 3 with jaundice [bilirubin 8.3, 11.9 and 13.4 mg/dL], one rechallenged with recurrence, no deaths, all recovering without transplantation). 28388864
Koller T, Galambosova M, Filakovska S, Kubincova M, Hlavaty T, Toth J, Krajcovicova A, et al. Drug-induced liver injury in inflammatory bowel disease: 1-year prospective observational study. World J Gastroenterol. 2017;23:4102-4111. (Among 251 patients with inflammatory bowel disease followed at a single referral center in Slovakia while monitoring for liver tests at 3 month intervals, ALT elevations above twice ULN arose in 3% but none above 5 times ULN and all were transient or due to other liver conditions while the combination of Alk P and GGT elevations arose in 1% but a higher proportion of those on azathioprine alone [3%] but none were associated with jaundice and only one required dose modification). 28652663
Wang CH, Chi MH, Lin JY, Chung WH, Chen CB. NUDT15 polymorphism identified in a patient with azathioprine hypersensitivity syndrome presenting as erythema nodosum and hepatotoxicity. Br J Dermatol. 2019;181:631-632.. (A 37 year old Chinese woman with idiopathic urticaria developed pruritus, fever, and rash two weeks after starting azathioprine [bilirubin 2.3 mg/dL, ALT 184 U/L, Alk P 184 U/L], skin biopsy demonstrating erythema nodosum and genetic analyses showing mutation in NUDT15, which is associated with excessive levels of thiopurine metabolites, especially in Asians). 30843183
Gisi K, Ispiroglu M, Kantarceken B, Sayar H. Severe cholestasis due to azathioprine in Behcet's disease. BMJ Case Rep. 2019;12:e226340. (33 year old Turkish man with Behcet disease developed pruritus and jaundice 1.5 months after starting azathioprine [bilirubin 18 mg/dL, ALT 57 U/L, Alk P 95 U/L, GGT 39 U/L, INR 1.6] improvement starting soon after stopping and all tests being normal 2 months later). 30936327
Kreijne JE, de Veer RC, de Boer NK, Dijkstra G, West R, Moorsel SAW, de Jong DJ, et al.; of the Dutch Initiative on Crohn, Colitis (ICC). Real-life study of safety of thiopurine-allopurinol combination therapy in inflammatory bowel disease: myelotoxicity and hepatotoxicity rarely affect maintenance treatment. Aliment Pharmacol Ther. 2019;50:407-415.. (Among 221 patients with inflammatory bowel disease treated with “low-dose thiopurine with allopurinol” in six medical centers in the Netherlands between 2009 and 2016, 34 patients initiated this approach because of hepatotoxicity, and it resolved in 29). 31359480
Nasser R, Kurnik D, Lurie Y, Nassar L, Yaacob A, Veitsman E, Waterman M, et al. Thiopurine hepatotoxicity can mimic intrahepatic cholestasis of pregnancy. Clin Res Hepatol Gastroenterol. 2020;44:e29-e31.. (31 year old Israeli woman with Crohn disease on long-term azathioprine continued therapy [75 mg daily] during a first pregnancy without difficulty but then required a dose increase to 125 mg daily and developed pruritus, rash, and abnormal liver tests during the 23rd week of a second pregnancy with persistence of symptoms and liver abnormalities (bilirubin 2.4 mg/dL, bile acids markedly elevated] despite ursodiol therapy but with prompt improvement on stopping azathioprine). 31109900
Roselli J, Innocenti T, Lynch EN, Parisio L, Macrì G, Milla M, Mello T, et al. Increased risk of liver cirrhosis during azathioprine therapy for Crohn's disease. Case Rep Gastrointest Med. 2020;2020:6726384. (49 year old man with long standing Crohn disease developed abnormal bilirubin after 3 years of azathioprine therapy [2 mg/kg/day] with bilirubin 2.2 mg/dL, ALT 26 U/L, Alk P 43 U/L,GGT 59 U/L, platelets 108,000/uL and biopsy said to demonstrate cirrhosis but is more compatible with nodular regenerative hyperplasia, laboratory features improving after stopping azathioprine). 32082651
Phillips J, Preskey R, Penfold C, Gordon F, Tyrrell-Price J. Liver steatosis is a risk factor for hepatotoxicity in inflammatory bowel disease patients treated with azathioprine. Eur J Gastroenterol Hepatol. 2020;32:1390-1394.. (Among 91 patients with inflammatory bowel disease treated with azathioprine, ALT levels increased more in those with steatosis by ultrasound before treatment [mean levels rising from 31 to 39 U/L than those without steatosis [mean levels changing from 19 to 18 U/L). 32091439
Schwartz B, Al-Sabti R, Reau N. Late-onset acute liver injury from azathioprine. ACG Case Rep J. 2022;9:e00847. (46 year old woman with chronic lymphocytic inflammation on azathioprine [150 mg twice daily] for 32 months presented with jaundice [bilirubin 4.3 rising to 8.8 mg/dL, ALT 95 rising to 127 U/L, Alk P 386 and later 89 U/L, INR 1.1 to 1.5], biopsy showing cholestatic hepatitis, and liver test abnormalities resolving rapidly once azathioprine was stopped). 36134121
Cataletti G, Santagata F, Pastorelli L, Battezzati PM. Severe azathioprine-induced liver injury 22 months after initiation of treatment. BMJ Case Rep. 2022;15:e253505. (50 year old woman with myasthenia gravis developed abdominal pain and jaundice 22 months after starting azathioprine at 300 mg daily [bilirubin 11.6 rising to 35.6 mg/dL, peak ALT 50 U/L, Alk P peak 222 U/L], with accompanying pancytopenia [platelets 27,000/μL, white count 1760/μL,Hgb 7.7 g/dL] and acute renal failure [creatinine 3.9 mg/dL] resolving completely with stopping and with normal tests 3 months later). 36543371
Chouchana L, Terris B, Sogni P, Treluyer JM, Costedoat-Chalumeau N, Loriot MA. Azathioprine-induced vanishing bile duct syndrome: The value of early thiopurine metabolism assessment. Br J Clin Pharmacol. 2023;89:2625-2630.. (34 year old woman with lupus erythematosus developed fluctuating aminotransferase elevations [ALT 150 and 115 U/L] 3 months after starting azathioprine [150 mg daily] and at 6 months developed jaundice and fatigue [bilirubin 4.9 mg/dL, ALT 46 U/L, Alk P 121 U/L] with high levels of methylmercaptopurine nucleotides [MMPN], low levels of 6-thioguanine nucleotides [6-TGN] and high thiopurine methyltransferase activity [TPMT]; liver test abnormalities persisted despite stopping therapy and liver biopsy showed bile duct paucity, whereafter liver tests slowly improved with time). 37218386
Frank Wolf M, Sloma R, Akria L, Rimon E, Wiener Y, Carmiel Haggai M, Lowenstein L. Azathioprine and 6-mercaptopurine-induced intrahepatic cholestasis of pregnancy: Case report and review of the literature. Taiwan J Obstet Gynecol. 2023;62:761-764.. (35 year old woman with Crohn disease and history of idiopathic cholestasis of pregnancy [ICP] on long-term mercaptopurine [50 mg/day] developed pruritus after 29 weeks of a 2nd pregnancy that worsened despite therapy with ursodiol, cholestyramine, and rifampin but improved rapidly with stopping mercaptopurine; identifies 11 cases of similar worsening of ICP with thiopurines ). 37679010
Makuuchi M, Kakuta Y, Umeno J, Fujii T, Takagawa T, Ibuka T, Miura M, et al.; Post-MENDEL study group; Kinouchi Y, Andoh A, Hisamatsu T, Masamune A. Real-world NUDT15 genotyping and thiopurine treatment optimization in inflammatory bowel disease: a multicenter study. J Gastroenterol. 2024;59:468-482. (Among 4628 Japanese adults with inflammatory bowel or Behcet’s disease treated with thiopurines with vs without prior genotyping for NUDT15 and dose adjustment, hepatotoxicity rates were not different [5.6% vs 5.1%] while severe leukopenia rates were less [0.7% vs 5.8%]). 38589597
Bentley BH, Cecil AE, Lippert WC. Atypical Intrahepatic cholestasis of pregnancy: a red herring. ACG Case Rep J. 2024;11:e01339. (20 year old pregnant woman on azathioprine and hydroxychloroquine for pulmonary hemosiderosis developed nausea and jaundice without pruritus at the 33rd week of gestation, the abnormalities resolving with spontaneous delivery and she later tolerated restarting azathioprine suggesting that the jaundice was due to idiopathic cholestasis of pregnancy). 38638198
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications including 7 attributed to azathioprine for an estimated incidence rate of 1 per 1,299 patients per year exposed). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 8 [2%] were attributed to azathioprine and 2 [0.9%] to mercaptopurine). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 17 cases [1.3%] attributed to azathioprine occurring at an estimated rate of 1 per 1:350 persons treated).
Dongre N, Kalita J, Misra UK. Azathioprine-induced veno-occlusive hepatotoxicity in a patient with myasthenia gravis. Curr Drug Saf. 2025;20:68-73.. (Abstract only: 35 year old man with myasthenia gravis treated with azathioprine for 5 years developed fatigue, abdominal pain, abnormal liver tests, and ultrasound findings suggestive of sinusoidal obstruction syndrome, which resolved after stopping azathioprine). 38265400
van Asseldonk DP, Crouwel F, Seinen ML, Scheffer PG, Veldkamp AI, de Boer NK, Lissenberg-Witte B, et al. Exploring the role of oxidative stress and the effect of N-acetylcysteine in thiopurine-induced liver injury in inflammatory bowel disease: a randomized crossover pilot study. Basic Clin Pharmacol Toxicol. 2024;134:507-518.. (Among 9 patients with inflammatory bowel disease and serum ALT elevations [less than 5 times ULN] during therapy with mercaptopurine [n=7] or azathioprine [n=2] who were continued on the thiopurine and given either N-acetylcysteine [1200 mg twice daily] or placebo for 4 weeks and then crossed-over to the alternative therapy, serum myeloperoxidase levels increased but there were no changes in the liver test abnormalities or levels of thiopurine metabolites). 38284479
Güven B, Yıldırım S, Aydın ZGG, İskenderoğlu GPR, Kamaşak T, Çakır M. Drug-induced liver injury in pediatric age group: Single-center experience. Pediatr Int. 2025;67:e70099.. (In a prospective database on drug-induced liver injury among admissions to a referral Turkish medical center between 2021 and 2023, 300 cases were enrolled attributed to 90 different drugs, mercaptopurine being the fifth most frequently implicated agent [n= 32, 5%], most cases being mild and 86% hepatocellular; azathioprine not listed among implicated agents). 40488674
Shi L, Wang Y, Qu Y, Chen R. Hepatotoxicity associated with anti-neoplastic agents: a pharmacovigilance analysis of the Food and Drug Administration Adverse Event Reporting System database. Front Immunol. 2025;16:1665425. (Analysis of reports of hepatotoxicity by antineoplastic agents made to the FDA’s Adverse Event Reporting System [FAERS] between 2004 and 2024 identified 4195 reports of the top 56 agents, mercaptopurine having the highest reporting odds ratio but only 67 reports compared to 766 for methotrexate, 306 rituximab, 245 pembrolizumab, and 188 nivolumab; azathioprine not listed). 41488639
Reinhart JM. Drug-induced liver injury. Vet Clin North Am Small Anim Pract. 2025;55:717-730. (Extensive review of drug-induced liver injury in veterinary animals mentions that cholestatic liver injury from azathioprine is dose related and arises in up to 15% of dogs but is rare in cats probably because of differences in concentrations of thiopurine methyltransferase). 40280782

## OTHER REFERENCE LINKS

1. Recent References on Azathioprine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Azathioprine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Azathioprine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Azathioprine)